# Methotrexate

## OVERVIEW

### Introduction

Methotrexate is an antineoplastic and immunosuppressive agent widely used in the therapy of leukemia, lymphoma, solid tumors, psoriasis and rheumatoid arthritis. When given in high intravenous doses, methotrexate can cause acute elevations in serum enzymes, and long term methotrexate therapy has been associated with frequent but mild elevations in serum liver enzymes and, more importantly, with development of chronic liver injury, progressive fibrosis, cirrhosis and portal hypertension.

### Background

Methotrexate (meth" oh trex' ate) is an antifolate and antimetabolite that is used extensively in the therapy of leukemia, lymphoma and several solid organ tumors. It also has potent immunomodulatory activity against psoriasis, inflammatory bowel disease and the inflammatory arthritidies. Methotrexate is considered a disease modifying antirheumatic drug (DMARD) and used widely in rheumatoid arthritis and other autoimmune diseases. Methotrexate acts by inhibition of folate metabolism, blocking dihydrofolic acid reductase, thereby inhibiting synthesis of purines and pyrimidines and decreasing DNA and RNA synthesis. Recent results suggest that methotrexate also leads to increase and release of adenosine, which may mediate its immunosuppressive activity. Folic acid antagonists (aminopterin) were developed in the late 1940s and introduced into clinical medicine shortly thereafter. Aminopterin was later replaced by methotrexate because of its better tolerance and lower rate of toxicity. Methotrexate was approved for use in cancer in the United States in 1955, for psoriasis in 1972 and rheumatoid arthritis in 1988 and is still widely used for these indications. Methotrexate is available in generic forms and under the brand names of Rheumatrex and Trexall in tablets of 2.5, 5, 7.5, 10 and 15 mg, and in both powdered and liquid-for-injection forms in vials of various strengths for intravenous, intramuscular or intrathecal injection. The dose regimen varies by indication; high, short term doses being used in treatment of cancer and chronic, lower doses for autoimmune conditions. The typical maintenance dose used to treat psoriasis and rheumatoid arthritis is 7.5 to 25 mg once weekly either orally or by injection. Side effects are mostly dose related and include stomatitis, oral ulcers, hair loss, fatigue, headache, gastrointestinal upset, nausea, diarrhea and bone marrow suppression. Severe adverse events include bone marrow suppression, severe infections, severe liver and lung disease, lymphomas, severe skin reactions, tumor lysis syndrome, fetal death and congenital abnormalities.

### Hepatotoxicity

Methotrexate is well known to cause serum aminotransferase elevations and long term therapy has been linked to development of fatty liver disease, fibrosis and even cirrhosis. The literature on methotrexate is extensive, but with great variability in rates of liver test and biopsy abnormalities at different doses, dose regimens and durations of therapy.

With high dose intravenous methotrexate, serum ALT levels can rise to 10 to 20 times the upper limit of normal (ULN) within 12 to 48 hours, but levels then fall rapidly to normal with only rare instances of jaundice or symptoms of liver injury. With long term, low-to-moderate dose methotrexate therapy, elevations in serum ALT or AST values occur in 15% to 50% of patients, but are usually mild and self-limiting. Approximately 5% of patients have elevations greater than twice normal and these abnormalities resolve rapidly with discontinuation or dose modification, but can resolve even with continuation at the same dose level. The reported rate of ALT elevations during therapy has varied considerably, perhaps because of differences in frequency of determinations (every month vs every 3, 6 or 12 months) and due to the timing of the blood sampling (whether just before or soon after the once weekly dose). Finally, coadministration of folic acid has been shown to decrease the frequency of serum enzyme elevations and now is commonly used.

Long term therapy with methotrexate has been associated with development of fatty liver and hepatic fibrosis and, in rare instances, portal hypertension and symptomatic cirrhosis. Symptoms are usually absent until cirrhosis is present, and liver tests are typically normal or minimally and transiently elevated. Routine monitoring of patients with regular liver biopsies done at 1 to 2 year intervals or with cumulative methotrexate doses of 1 to 10 grams demonstrates that approximately 30% of patients develop mild-to-moderate histological abnormalities (fat, cellular unrest, mild inflammation, nuclear atypical) and 2 to 20% of patients develop some degree of hepatic fibrosis. Well documented cases of cirrhosis arising during long term methotrexate therapy have been reported, but cirrhosis is rare in prospective series, even with routine histological monitoring. Patients who develop fibrosis on long term methotrexate therapy often have other risk factors for fatty liver disease, including excessive alcohol use, obesity, diabetes and concurrent administration of other potentially hepatotoxic agents. Use of high doses and daily methotrexate dosing is particularly associated with development of hepatic fibrosis and rates of cirrhosis of greater than 20% after 5 to 10 years of treatment. With more modern dose regimens (5 to 15 mg in one dose weekly with folate supplementation), fibrosis and clinically apparent liver disease are rare even with long term use. The hepatic fibrosis and cirrhosis due to methotrexate typically arise after 2 to 10 years of treatment and can present with ascites, variceal hemorrhage or hepatosplenomegaly. Some patients present with signs and symptoms of portal hypertension, yet have only moderate degrees of fibrosis, suggesting that methotrexate may also cause nodular regeneration. Patients who develop portal hypertension and cirrhosis usually have had minimal or no elevations in serum aminotransferase or alkaline phosphatase levels, and monitoring using serum enzymes appears to be poorly predictive of fibrosis development. Noninvasive markers of hepatic fibrosis, such as serial platelet counts, serum procollagen III aminoterminal peptide (PIIIP), serum bile acids, hepatic ultrasound, advanced imaging techniques and transient elastography may be more efficient in screening for fibrosis in patients on long term methotrexate, but the reliability and accuracy of these approaches has not been documented prospectively. Patients with cirrhosis due to methotrexate are often asymptomatic and the condition tends to be non-progressive, even in those who restart low dose therapy. Rare instances of hepatocellular carcinoma have been reported in patients with suspected methotrexate induced cirrhosis.

Low dose, long term methotrexate therapy has also been implicated in rare instances of reactivation of hepatitis B in patients with rheumatoid arthritis or psoriasis who were HBsAg carriers, without HBeAg and with normal ALT levels and no detectable or low levels of HBV DNA before starting methotrexate. The frequency of reactivation with methotrexate is unknown, but is probably low. Reactivation typically presents after years of therapy with methotrexate and most published cases were also receiving corticosteroids. The clinical presentation is characterized by insidious onset of fatigue, nausea and jaundice accompanied by marked elevations in serum ALT and HBV DNA levels. In some instances, the acute injury is severe and progressive resulting in liver failure. In many case reports, reactivation occurred when methotrexate was withdrawn, perhaps as a result of restoration of immune reactivity in those in whom HBV DNA levels have risen during treatment. Reactivation has also been described in patients with antibodies to HBV without HBsAg (reverse seroconversion) treated with methotrexate and prednisone. The cases of reactivation of hepatitis B published in the literature have mostly resulted in death or emergency liver transplantation, perhaps reflecting publication bias for more severe cases. These cases have led to recommendations for routine screening for HBsAg before starting long term methotrexate therapy and prophylaxis with antiviral agents or careful monitoring for rises in HBV DNA levels if methotrexate is used. However, whether methotrexate on its own, without prednisone, can cause reactivation of hepatitis B is not clear.

Likelihood score: A (well known cause of chronic, clinically significant liver injury, portal hypertension and cirrhosis).

### Mechanism of Injury

The mechanism of liver injury with methotrexate is believed to be direct toxicity, through inhibition of RNA and DNA synthesis in the liver and producing cellular arrest. Methotrexate therapy has been shown to increase hepatic stellate cell numbers, but the mechanism by which fibrosis is induced has not been clearly elucidated. Concurrent therapy with folate has been shown to reduce the rate of serum enzyme elevations during low dose methotrexate therapy.

### Outcome and Management

Methotrexate can lead to serious liver disease, portal hypertension, fibrosis and cirrhosis, usually with long term use particularly when given in daily regimens and in higher doses. Various guidelines have been developed and refined for monitoring of patients with psoriasis or rheumatic disorders during long term methotrexate use, although the effectiveness and necessity of these approaches are often debated. At present, both the American Academy of Dermatology and the American College of Rheumatology recommend careful evaluation of patients before initiating methotrexate therapy for evidence of liver disease and risk factors for developing fatty liver. While a pretreatment liver biopsy is no longer recommended for all patients, a biopsy is recommended in patients with any evidence of liver disease or significant risk factor (excessive alcohol use, chronic viral hepatitis, elevations in serum enzymes, and in selected patients with diabetes and obesity). Patients should be told to avoid alcohol use, and abstinence is often recommended. Concurrent administration of folic acid (~1 mg daily) has been shown to decrease the rate of liver test abnormalities on therapy without apparently affecting the efficacy of methotrexate. On-treatment monitoring of serum aminotransferase levels is recommended on a monthly basis for at least 6 months and then every 3 months, with more intensive monitoring and withdrawal of therapy if aminotransferase levels rise and stay above 3 times the ULN. Routine liver biopsy after a cumulative dose of 1, 3 and 8 grams of methotrexate is considered prudent, but guidelines from different societies vary on this issue. Alternatively, monthly aminotransferase levels can be monitored and patients with raised values at least 50% of the time might be candidates for surveillance liver biopsy. A system for grading of liver biopsies has been developed and widely used (Roenigk Scale). Patients with Roenigk IIIb (advanced fibrosis) or IV (cirrhosis) are advised to stop therapy. With improvement in noninvasive tests for liver fibrosis such as transient elastography and serum fibrosis markers, recommendations for surveillance liver biopsies will undoubtedly be relaxed. There does not appear to be cross reactivity in hepatic side effects between methotrexate and other disease modifying antirheumatic drugs (DMARDs) such as leflunomide, hydroxychloroquine, azathioprine, etanercept, or infliximab.

Drug Class: Antineoplastic Agents; Antirheumatic Agents; Dermatologic Agents; Gastrointestinal Agents

## CASE REPORTS

### Case 1. Cirrhosis and ascites after long term therapy with methotrexate.(1)

A 38 year old woman with rheumatoid arthritis who had been treated with prednisone, d-penicillamine and gold was switched to methotrexate (7.5 mg/week) and salicylate (3.9 g/day) because of poor response to the other agents. Her serum enzymes and bilirubin levels were normal and serum albumin 3.7 g/dL. Her arthritis symptoms improved on methotrexate therapy, and the dose was raised to 15 mg/week. After two years of methotrexate therapy, she underwent a routine surveillance liver biopsy which showed changes of steatosis and mild portal inflammation (Roenigk grade 1). Serum AST and alkaline phosphatase were still normal, but albumin levels had decreased to 3.2 g/dL. One year later, a repeat surveillance liver biopsy showed mild fibrosis and steatosis (Roenigk grade IIIA). A third liver biopsy done after 4 years of therapy (total dose 2.2 g) again showed moderate activity, steatosis and mild fibrosis. Serum aminotransferase and alkaline phosphatase levels were normal. One year later (year 5 of therapy), she presented with weight gain, peripheral edema and ascites. Serum ALT was 17 U/L, AST 35 U/L, bilirubin 0.2 mg/dL, albumin 2.4 g/dL and prothrombin time 18.4 seconds. She denied alcohol use or previous history of liver disease or exposures to viral hepatitis. Tests for hepatitis A and B were negative as were routine autoantibodies. A liver biopsy showed bridging fibrosis and moderate inflammation (Roenigk grade IIIB), but not frank cirrhosis. Methotrexate and salicylate were stopped and she improved clinically with resolution of the peripheral edema and ascites. Serum albumin levels rose and prothrombin time fell into the normal range. She was later maintained on salicylate alone.

#### Key Points

Medication: | Methotrexate (15 mg/week) for 5 years
Pattern: | Undefined (minimal or no serum enzyme elevation)
Severity: | 4+ (ascites)
Latency: | 5 years
Recovery: | Clinical improvements over the ensuing 4-6 months
Other medications: | Salicylate 3.9 g/day, prednisone 7.5 mg/day

#### Comment

Long term, low dose methotrexate is associated with insidious development of hepatic fibrosis in at least 5% of patients, which in some instances leads to cirrhosis and liver decompensation. The absence of serum enzyme elevations accompanying this progressive fibrosis makes it difficult to monitor patients short of performing routine surveillance liver biopsies at 1 to 2 year intervals. As shown in this example, even surveillance liver biopsies may not adequately reflect the severity of the liver injury and allow for stopping therapy before onset of serious fibrosis. Somewhat typical of fibrotic liver injury caused by methotrexate was the lack of accompanying clinical symptoms and the clinical improvement that occurred when methotrexate was stopped. The fact that the liver biopsy did not show frank cirrhosis, suggests that the portal hypertension may have been due in part to nodular regeneration. Salicylates decrease renal elimination of methotrexate and displace methotrexate from protein binding, and thus may increase the likelihood of toxicity.

### Case 2. Cirrhosis after long term therapy with methotrexate.(2)

A 51 year old man with active rheumatoid arthritis was treated with methotrexate at an initial dose of 7.5 mg weekly, increasing to 15 mg weekly with daily folic acid and low doses of prednisone (5 mg daily) for four years with only partial control of his arthritis. He was then enrolled in an open label trial of the combination of methotrexate and leflunomide (10 mg/day). He had significant improvement and continued on both drugs for a total of 3.5 years. During the first year of therapy, he had minor and transient serum ALT elevations, but none were more than 3 times the upper limit of normal (ULN) (Table). Six months into combination therapy, however, his platelet count began to fall, and it remained low despite a decrease in the dose of methotrexate to 5 mg weekly. After 3.5 years of combination therapy, an abdominal ultrasound showed mild hepatomegaly, splenomegaly with increased echogenicity of the liver suggestive of fatty infiltration. He denied alcohol use and any history or risk factors for liver disease. He had been treated with methotrexate for 7.5 years and received a cumulative dose of 4.5 g. Tests for hepatitis A, B and C were negative as were routine autoantibody tests. Liver tests including serum aminotransferase levels, alkaline phosphatase, bilirubin and albumin were normal and prothrombin time was not increased. A percutaneous liver biopsy showed marked fibrosis, early cirrhosis, mild steatosis and nuclear variability without inflammation or obvious necrosis.

#### Key Points

Medication: | Methotrexate (5-15 mg/week) for 7.5 years (total dose 4.5 g)
Pattern: | Undefined (no serum enzyme elevation)
Severity: | 4+ (cirrhosis)
Latency: | ~5 years
Recovery: | Not mentioned
Other medications: | Leflunomide (10 mg/day for 3 years), folic acid, prednisone (5 mg/day)

#### Laboratory Values

Years After Starting | ALT (U/L) | Alk P (U/L) | Platelets (per μL) | Other
4.0 | 38 | 101 | 181,000 | Leflunomide started
4.2 | 39 | 119 | 206,000
4.4 | 57 | 111 | 150,000
4.6 | 28 | 105 | 129,000
4.8 | 27 | 111 | 109,000
5.0 | 38 | 106 | 105,000 | Methotrexate dose reduced
5.5 | 37 | 117 | 98,000
6.0 | 32 | 107 | 103,000
6.5 | 28 | 101 | 96,000
7.0 | 73 | 109 | 92,000 | Bilirubin and albumin normal
7.5 | 21 | 115 | 148,000 | Liver biopsy
Normal | <44 | <111 | >160,000

#### Comment

This case demonstrates how significant hepatic fibrosis and portal hypertension can arise during methotrexate therapy without accompanying symptoms or significant elevations in serum aminotransferase levels. Also characteristic was the mild and nonprogressive nature of the cirrhosis despite continuation of methotrexate. A possible noninvasive marker for the development of significant fibrosis in this case was the decrease in platelet count, which fell from 181,000/μL at baseline to 105,000 μ/L one year later–a 47% decline and a “platelet slope” of -74,000/year. In analyses of serial platelet count determinations in patients who developed portal hypertension, a platelet slope of -9,000/year was found to be indicative of the development of portal hypertension and hepatic dysfunction. Whether leflunomide contributed to the toxicity of methotrexate is not clear, but the findings are compatible with methotrexate toxicity based upon the duration and total dose received. The patient did not have typical risk factors for developing methotrexate related fibrosis such as excessive alcohol use, underlying viral hepatitis, renal insufficiency or diabetes (no mention is made of body weight or presence of obesity). While this patient did not qualify for undergoing surveillance liver biopsies (according to the criteria of the American College of Rheumatology), noninvasive tests such as PIIIP, hepatic imaging or elastography would have been appropriate and would likely have suggested the presence of significant fibrosis much earlier.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Methotrexate – Generic, Trexall®

DRUG CLASS

Antineoplastic Agents

Antirheumatic Agents

Dermatologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=METHOTREXATE)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Methotrexate | 59-05-2 | C20-H22-N8-O5

## CITED REFERENCES

1 Clegg DO, Furst DE, Tolman KG, Pogue R. (1989). Acute, reversible hepatic failure associated with methotrexate treatment of rheumatoid arthritis. J Rheumatol.
2 Weinblatt ME, Dixon JA, Falchuk KR. (2000). Serious liver disease in a patient receiving methotrexate and leflunomide. Arthritis Rheum.

## ANNOTATED BIBLIOGRAPHY

References updated: 19 February 2020

Zimmerman HJ. Methotrexate. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 681-7. (Expert review of hepatotoxicity of methotrexate published in 1999).
Aithal GP. Hepatotoxicity related to methotrexate. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 593-604. (Review of clinical features, course and outcome of methotrexate hepatotoxicity with discussion and comparison of guidelines for monitoring).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Antimetabolites. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1177-80. (Textbook of pharmacology and therapeutics).
Colsky J, Greenspan EM, Warren TN. (1955). Hepatic fibrosis in children with acute leukemia after therapy with folic acid antagonists. AMA Arch Pathol. (Five children with acute leukemia who had remission with aminopterin or methotrexate therapy developed cirrhosis within 8 months to 1.5 years of starting therapy).
Hutter RVP, Shipkey FH, Tan CTC, Murphy ML, Chowdhury M. (1960). Hepatic fibrosis in children with acute leukaemia: a complication of therapy. Cancer. (Review of liver histology from autopsies on 273 children with leukemia; rate of fibrosis increased with introduction of chemotherapy, including antifolates aminopterin and methotrexate from 31% [usually mild] to 84% [29% moderate and 1% severe]).
Ryan TJ, Vickers HR, Salem SN, Callender ST, Badenoch J. (1964). The treatment of psoriasis with folic acid antagonists. Br J Dermatol. (Among 14 patients with psoriasis treated with aminopterin or methotrexate using a daily schedule and rest periods, 4 had elevations in ALT [62-122 U/L], rapidly returning to normal upon stopping; liver biopsy in one patient showed steatosis).
O’Rourke RA, Eckert GE. (1964). Methotrexate-induced hepatic injury in an adult. A case report. Arch Intern Med. (62 year old with psoriasis treated with methotrexate for 2 years [25-50 mg/week] had AST 66 U/L, Alk P 1.5 times ULN, bilirubin 0.6 mg/dL, and liver biopsy showing mild fatty change and periportal fibrosis).
Taft LI. (1965). Methotrexate induced hepatitis in childhood leukemia. Isr J Med Sci. (Among 32 Australian children with acute leukemia treated with methotrexate for more than a month, 7 developed evidence of cirrhosis [ascites in 6, jaundice in 1] which was documented by liver biopsy in 3; after only 3-10 months of therapy, improving clinically with stopping therapy).
Hersh EM, Wong VG, Henderson ES, Freireich EJ. (1966). Hepatotoxic effects of methotrexate. Cancer. (Analysis of 22 patients given high doses of methotrexate [2-4 five-day courses at 10-22 mg/m^2^], ALT levels rose in ~90% of patients, peak levels of 37-1100 U/L, resolving with stopping therapy; biopsies in 12 patients showed portal inflammation in 6, fatty change in 5, fibrosis in 1).
Talerman A, Thompson RB. (1966). Hepatic fibrosis in a child possibly due to prolonged methotrexate. J Clin Pathol. (11 year old child with leukemia treated with methotrexate for 3 years [total dose 2.5 g] died of leukemic relapse and had hepatomegaly with extensive hepatic fibrosis and steatosis on autopsy).
Fry L. (1966). The treatment of psoriasis with parenteral methotrexate. Br J Dermatol. (Among 15 patients treated for psoriasis with weekly parenteral methotrexate doses of 25-100 mg for 1-6 months, 9 developed raised AST levels [58-208 U/L], usually lasting for less than 7 days after an injection, all resolving with stopping).
Coe RO, Bull FE. (1968). Cirrhosis associated with methotrexate treatment of psoriasis. JAMA. (Three patients developed cirrhosis during methotrexate therapy for psoriasis with insidious onset after 1, 2 and 5.5 years with minimal elevations in ALT [peak 53-132 U/L], Alk P [1.2-2 times ULN], and bilirubin [0.9-1.9 mg/dL], presenting with peripheral edema, ascites and hepatomegaly).
Auerbach R. (1969). Cirrhosis and methotrexate treatment of psoriasis. JAMA. (Letter in response to Coe and Bull questioning relationship of liver injury and methotrexate).
Roenigk HH, Fowler-Bergfeld W, Curtis GH. (1969). Methotrexate for psoriasis in weekly oral doses. Arch Dermatol. (Among 204 patients with psoriasis treated with oral methotrexate [25 mg weekly], AST elevations occurred in 6.8%, but liver biopsies done on patients with abnormal liver tests found "no significant pathologic changes").
Dahl MG. (1969). Methotrexate and the liver. Br J Dermatol. (Description of 3 patients who developed hepatic fibrosis on oral methotrexate for psoriasis for up to 2.5 years).
Dubin HV, Harrell ER. (1969). Absorption of methotrexate and hepatotoxicity. JAMA. (Letter in response to Baker and Dahl raising issue of variability in absorption of methotrexate as basis for variability in rates of hepatotoxicity).
Epstein EH, Croft JD. (1969). Cirrhosis following methotrexate administration for psoriasis. Arch Dermatol. (46 year old man with psoriasis developed cirrhosis after 5 years of methotrexate therapy [10-80 mg/week] with jaundice, [bilirubin 7.4 mg/dL, ALT 35 U/L, Alk P 1.5 times ULN], ascites and hepatomegaly, dying 4 months later of end stage liver disease and autopsy showing small nodular liver with diffuse fibrosis and fatty change).
McDonald CJ, Bertino JR. (1969). Parenteral methotrexate in psoriasis. A report on the efficacy and toxicity of long-term intermittent treatment. Arch Dermatol. (Results of methotrexate therapy in 36 patients with psoriasis; side effects included elevations in AST in 4 patients, 2 of whom had cirrhosis, but both were alcoholic and improved with stopping alcohol intake).
Muller SA, Farrow GM, Martalock DL. (1969). Cirrhosis caused by methotrexate in the treatment of psoriasis. Arch Dermatol. (Two cases of cirrhosis arising in patients with psoriasis on methotrexate; 37 and 52 year old men treated for 7 and 5 years with normal AST levels and improvement on stopping therapy).
Sharp H, Nesbit M, White J, Krivit W. (1969). Methotrexate liver toxicity. J Pediatr. (Prospective study of 10 children receiving methotrexate [7 on daily and 4 on intermittent therapy for leukemia] found hepatic fibrosis and fat even without liver test abnormalities, often improving after stopping therapy).
(1970). Psoriasis, methotrexate, and cirrhosis. JAMA. (Editorial recommending caution in using methotrexate particularly because "results of liver-function tests may be deceiving because transient abnormalities frequently occur in the absence of significant hepatotoxicity, while irreversible liver damage may exist despite normal results").
Bender AS. (1970). Hazards of prolonged low-dose methotrexate therapy. Va Med Mon.
Dubin HV, Harrell ER. (1970). Liver disease associated with methotrexate treatment of psoriatic patients. Arch Dermatol. (Three men with psoriasis, ages 23, 41 and 51 years, treated with methotrexate for 2-8 years had liver biopsies showing fibrosis, ballooning degeneration and inflammation, with poor correlation to AST elevations which were intermittent and mild).
Holst R, Mobacken H. (1970). Nord Med. (Three patients with psoriasis on methotrexate had abnormal liver biopsy findings of inflammation and steatosis).
Weinstein GD, Cox JW, Suringa DW, Millard MM, Kalser M, Frost P. (1970). Evaluation of possible chronic hepatotoxicity from methotrexate for psoriasis. Arch Dermatol. (Analysis of liver biopsies done on 29 patients with psoriasis; among 21 on methotrexate, 16 had steatosis, 2 had fibrosis and 1 cirrhosis [78 year old woman treated for 2 years]; among 8 on no therapy 4 had steatosis but none had fibrosis and all had normal ALT and AST levels).
Almeyda J, Baker H, Levene GM, Barnardo D, Landells JW. (1971). Methotrexate, alcohol, and liver damage. Br Med J. (Among 39 patients with psoriasis on methotrexate undergoing liver biopsy, 12 had fibrosis and 3 cirrhosis [all 3 were heavy drinkers]; among 20 patients not on methotrexate, 3 had fibrosis).
Almeyda J, Barnardo D, Baker H. (1971). Drug reactions XV. Methotrexate, psoriasis and the liver. Br J Dermatol. (Review of hepatotoxicity of methotrexate in psoriasis based upon 7 publications; among 130 biopsies done before therapy 29% were normal, 57% had mild or nonspecific changes, 5% fibrosis and 1.5% cirrhosis often corresponding to alcohol history; among 193 biopsies done during methotrexate therapy, 21% were normal, 23% had fibrosis and 11% cirrhosis, with marked variability in rates of cirrhosis [5-16%]; alcohol could not explain all hepatic fibrosis associated with methotrexate therapy).
Baker H. (1971). Liver damage and methotrexate. Br Med J. (Comments on drug levels with daily versus weekly dosing of methotrexate).
Dahl MG, Gregory MM, Scheuer PJ. (1971). Liver damage due to methotrexate in patients with psoriasis. Br Med J. (Among 37 patients with psoriasis treated with methotrexate who were not heavy drinkers, cirrhosis was present in 7 [19%], fibrosis in 10 [27%] and minor abnormalities in 17 [46%] including fat, ballooning degeneration and inflammation; fibrosis appeared only after 10 months and correlated with duration of therapy; nonspecific findings of fat and inflammation can be seen in pretreatment biopsies; AST elevations occurred in almost all patients, but were mild and transient and did not predict the severity of biopsy changes).
Filip DJ, Logue GL, Harle TS, Farrar WH. (1971). Pulmonary and hepatic complications of methotrexate therapy of psoriasis. JAMA. (49 year old man with psoriasis developed pulmonary toxicity and liver disease [biopsy showing fat and fibrosis] after 5 years of methotrexate therapy, improving on withdrawal).
Price LA. (1971). Liver damage and methotrexate. Br Med J. (Letter arguing for use of folinic acid when using methotrexate even in oral low dose therapy).
Roenigk HH, Bergfeld WF, St Jacques R, Owens FJ, Hawk WA. (1971). Hepatotoxicity of methotrexate in the treatment of psoriasis. Arch Dermatol. (Liver biopsies in 50 patients with psoriasis; 7 of 13 had abnormal histology before therapy which correlated with alcohol history; 28 of 37 taken during methotrexate therapy were abnormal including 6 with cirrhosis; initial scoring system proposed with 1=normal; 2=minor steatosis; 3=moderate-to-severe steatosis and inflammation; 4=fibrosis; 5=cirrhosis).
Tashima CK. (1971). Methotrexate and hepatic disease. JAMA. (70 year old woman with psoriasis presented with cirrhosis and end stage liver disease after being treated with methotrexate for 4 years; alcohol history unclear).
Vogler WR, Jacobs J. (1971). Toxic and therapeutic effects of methotrexate-folinic acid(Leucovorin) in advanced cancer and leukemia. Cancer. (Toxicity of high dose methotrexate followed by leucovorin rescue in patients with cancer and leukemia; little on hepatotoxicity).
Zachariae H, Schiodt T. (1971). Liver biopsy in methotrexate treatment. Acta Derm Venereol. (Analysis of 57 liver biopsies from 36 patients with psoriasis on methotrexate therapy showed high rate of findings in pretreatment biopsies and no significant change except for increase in steatosis on treatment; ALT elevations occurred but liver biopsies often showed no abnormalities; no mention of fibrosis).
Almeyda J, Barnardo D, Baker H, Levene GM, Landells JW. (1972). Structural and functional abnormalities of the liver in psoriasis before and during methotrexate therapy. Br J Dermatol. (Liver biopsies on 67 patients with psoriasis comparing 25 not on therapy to 42 on methotrexate [for 0.3-7 years]: 56% vs 40% were normal, 28% vs 24% had nonspecific, mild changes, 16% vs 29% had fibrosis and 0% vs 7% had cirrhosis; fibrosis more common with daily dose regimens and in alcoholics).
Dahl MG, Gregory MM, Scheuer PJ. (1972). Methotrexate hepatotoxicity in psoriasis--comparison of different dose regimens. Br Med J. (Analysis of liver biopsies from 44 patients with psoriasis treated with methotrexate, found 6 with cirrhosis [13%] and 11 fibrosis [25%]; presence of fibrosis correlating with duration of therapy and with daily [12 of 22] rather than weekly [2 of 14] dosing).
Griesman FA, Hammer CJ, Fenster LF. (1972). Methotrexate-associated liver disease in psoriatic patients. Northwest Med.
Ryan TJ, Sadler GH, Guerrier C, Vickers HR. (1972). Methotrexate hepatotoxicity in psoriasis. Br Med J. (Among 4 patients with psoriasis on methotrexate for more than 10 years using daily regimens, 2 had cirrhosis, but 2 had no fibrosis on biopsy).
Robeson JA, Spenney J, Hirschowitz BI. (1972). Cirrhosis following prolonged treatment of psoriasis with methotrexate orally. South Med J. (60 year old non-drinking woman with psoriasis on methotrexate for 9 years presented with cirrhosis and ascites [bilirubin 1.0 mg/dL, AST 25, Alk P 2.5 times ULN, albumin 2.7, prothrombin index 63]; patient improved clinically on withdrawal).
Roenigk HH, Maibach HI, Weinstein GD. (1972). Use of methotrexate in psoriasis. Arch Dermatol. (Recommended liver biopsy before starting methotrexate and repeat liver biopsy based upon abnormal liver tests and proposed a five-point grading system from normal [Grade I] to cirrhosis [Grade 5]).
Roenigk HH, Maibach HI, Weinstein GP. (1973). Methotrexate therapy for psoriasis. Guideline revisions. Arch Dermatol. (Change in grading system to: Grade I=normal or mild fatty infiltration, nuclear variability and portal inflammation; II=moderate changes; III=fibrosis [with septa]; IV=cirrhosis; with recommendations not to use or continue methotrexate in patients with Grade III changes and to perform a liver biopsy before starting therapy).
Weinstein G, Roenigk H, Maibach H, Cosmides J, Halprin K, Millard M, et al. (1973). Psoriasis-liver-methotrexate interactions. Arch Dermatol. (Cooperative study with analysis of 742 biopsies from 550 patients with psoriasis on methotrexate from 10 clinical centers; ALT levels elevated in 12% before and 13% after methotrexate; moderate-severe fibrosis in 7% vs 13%, cirrhosis in 1.5% vs 2.6%, fibrosis correlating with duration and cumulative dose, daily dosing, alcohol intake, obesity and diabetes).
Coughlin GP, Henderson DW, Reid JG, Grant AK. (1973). Cirrhosis following methotrexate administration for psoriasis. Med J Aust. (52 year old with psoriasis [non-drinker] treated with methotrexate [daily regimens] for 3 years presented with large liver, AST 50 U/L, Alk P 1.5 times ULN, albumin 30 gm/dL, platelets 37,000/μL, and biopsy showing cirrhosis; improved clinically upon withdrawal).
Horvath E, Kovacs K, Ross RC. (1973). Liver ultrastructure in methotrexate treatment of psoriasis. Arch Dermatol. (Analysis of 9 biopsies from patients with psoriasis on methotrexate which had only mild, nonspecific changes on light microscopy but showed increase in Ito cells by electron microscopy).
Kraus Z, Vortel V, Fixa B, Komárková O. (1973). Cesk Dermatol.
Moldenhauer E, Dabels J, Diwok K, Leithäer W, Nowotny P. (1973). Dermatol Monatsschr.
Pai SH, Werthamer S, Zak FG. (1973). Severe liver damage caused by treatment of psoriasis with methotrexate. N Y State J Med. (32 year old with psoriasis treated with methotrexate for 3 years [0.5 g] presented with fever, coma and acidosis; autopsy showed advanced fibrosis; no liver tests or alcohol history provided).
Palmer HM. (1973). Hepatotoxicity of methotrexate in the treatment of psoriasis. Practitioner. (Analysis of 37 patients with psoriasis on long term methotrexate, usually 5 days a week for 2 months to 6 years; 4 of 23 biopsies showed fibrosis and 3 cirrhosis [after 1.8-2.8 g total dose]).
Podurgiel BJ, McGill DB, Ludwig J, Taylor WF, Muller SA. (1973). Liver injury associated with methotrexate therapy for psoriasis. Mayo Clin Proc. (Among 35 patients with psoriasis treated with methotrexate for 1 to 8 years, liver biopsies showed fibrosis in 5 [14%] and cirrhosis in 4 [11%]; presence of fibrosis correlated with AST elevations, >2 years of therapy, and daily administration).
Tobias H, Auerbach R. (1973). Hepatotoxicity of long-term methotrexate therapy for psoriasis. Arch Intern Med. (Liver biopsy results on 88 patients with psoriasis treated with methotrexate found increase in fibrosis and cirrhosis after cumulative dose of 2 g; rates higher in alcoholics; fat was present in 64% of 14 untreated versus 61% of 41 treated non-users of alcohol; nuclear changes found in most treated patients; ALT and AST usually normal).
Millward-Sadler GH, Ryan TJ. (1974). Methotrexate induced liver disease in psoriasis. Br J Dermatol. (Among 19 patients with psoriasis treated with methotrexate for 1-10 years, 2 had fibrosis and 3 cirrhosis; fibrosis correlated with duration of therapy and was more common with daily vs weekly regimens; serum liver tests were not helpful in identifying patients with fibrosis).
Reese LT, Grisham JW, Aach RD, Eisen AZ. (1974). Effects of methotrexate on the liver in psoriasis. J Invest Dermatol. (Among 102 liver biopsies done in 70 patients with psoriasis, fibrosis was present in 1 of 35 [3%] untreated versus 3 of 35 [9%] on methotrexate [1 with cirrhosis], but nonspecific changes were found equally in the two groups, and serum enzyme elevations did not correlate with histological findings).
Ruszczak Z, Prószynska-Kuczynska W, Krajewski C. (1974). Wiad Lek.
Shapiro HA, Trowbridge JO, Lee JC, Maibach HI. (1974). Liver disease in psoriatics - an effect of methotrexate therapy?. Arch Dermatol. (Among 67 patients with psoriasis, liver fibrosis and fat did not correspond with methotrexate therapy; cirrhosis present in 4 of 20 [20%] before therapy and 5 of 46 [12%] on methotrexate; amount of fat and liver tests abnormalities were also similar in untreated and treated patients).
Delbrück H, Schaison G, Chelloul N, Bernard J. (1975). Dtsch Med Wochenschr. (12 year old girl on maintenance methotrexate and mercaptopurine for 7 years after remission in acute leukemia presented with hepatocellular carcinoma).
Warin AP, Landells JW, Levene GM, Baker H. (1975). A prospective study of the effects of weekly oral methotrexate on liver biopsy. Br J Dermatol. (25 patients with psoriasis underwent 192 liver biopsies before and after 1-5 years of weekly oral methotrexate therapy showed no increase in fibrosis or inflammation; pretreatment liver biopsies in 66 patients were normal in 67%, had nonspecific changes in 26%, fibrosis in 6% and cirrhosis in 1 alcoholic patient).
Nyfors A, Svejgaard A. (1976). The relation of HL-A antigens to liver histology in methotrexate-treated psoriatics. Acta Derm Venereol. (In 45 patients with psoriasis on methotrexate therapy [14 with cirrhosis or fibrosis], no association was found between HLA-A and liver histological findings).
Hopwood D, Nyfors A. (1976). Effect of methotrexate therapy in psoriatics on the Ito cells in liver biopsies, assessed by point-counting. J Clin Pathol. (Among 24 patients with psoriasis treated with methotrexate, light and electron microscopy of liver tissue showed increase in hepatic stellate cells [mean volume density rising from 0.25% to 0.66%] with methotrexate therapy, not correlating with dose and decreasing rapidly with stopping; morphology of stellate cells did not change).
Nyfors A, Poulsen H. (1976). Liver biopsies from psoriatics related to methotrexate therapy. 1. Findings in 123 consecutive non-methotrexate treated patients. Acta Pathol Microbiol Scand A. (Among 123 liver biopsies in patients with psoriasis not on methotrexate, 49% were normal, 37% had fatty change, 12% had nonspecific findings, 1% fibrosis and 1% cirrhosis; abnormalities correlating with raised AST [high specificity, low sensitivity], alcohol history, age and obesity).
Nyfors A, Poulsen H. (1976). Liver biopsies from psoriatics related to methotrexate therapy. 2. Findings before and after methotrexate therapy in 88 patients. A blind study. Acta Pathol Microbiol Scand A. (Among 88 patients with psoriasis undergoing liver biopsy before and after 2-72 months [175-4590 mg] of weekly doses of methotrexate, 6 [7%] developed cirrhosis and 5 [6%] fibrosis with little correlation with dose, alcohol history, AST elevations or pretreatment liver histology).
Nyfors A. (1977). Liver biopsies from psoriatics related to methotrexate therapy. 3. Findings in post-methotrexate liver biopsies from 160 psoriatics. Acta Pathol Microbiol Scand A. (Among 160 patients with psoriasis treated with methotrexate, 92 had a single liver biopsy on therapy of whom 1% had cirrhosis and 7% fibrosis [correlated with alcohol intake and age but not total dose]; among 68 with two liver biopsies on therapy [total dose 175-5568 mg], 21% had cirrhosis and 24% fibrosis, fibrosis correlating with alcohol intake during therapy, obesity and older age, but cirrhosis found almost only in patients with >2 g methotrexate exposure).
Nyfors A, Hopwood D. (1977). Liver ultrastructure in psoriatics related to methotrexate therapy. 1. A prospective study of findings in hepatocytes from 24 patients before and after methotrexate treatment. Acta Pathol Microbiol Scand A. (Liver biopsies taken before and during methotrexate therapy in 24 patients with psoriasis showed increase in hepatocyte membrane whorls and vacuoles and increase in autophagic vacuoles, but no correlation with duration of therapy or total dose).
Hopwood D, Nyfors A. (1977). Liver ultrastructure in psoriatics related to methotrexate therapy. 2. Findings in bile ducts from 11 methotrexate treated psoriatics and 2 controls. Acta Pathol Microbiol Scand A. (Bile duct histology was studied by light and electron microscopy in 11 patients with psoriasis on methotrexate and 2 controls showed increase in autophagic vacuoles in biliary epithelial cells and nonspecific findings of mitochondrial damage and membrane whorls and particulate debris in lumen).
Horvath E, Kovacs K, Ross RC, Saibil F, Kerenyi NA. (1977). Desmosomal abnormalities in the liver of methotrexate-treated psoriatics. Experientia. (Among 50 liver biopsies from patients with psoriasis on methotrexate for 0.1 to 15 years, detachment of desmosomes was found in half of cases along with microfilaments anchored to mitochondria).
Nyfors A, Poulsen H. (1977). Morphogenesis of fibrosis and cirrhosis in methotrexate-treated patients with psoriasis. Am J Surg Pathol. (Analysis of progression of fibrosis using 31 liver biopsies from 8 patients with psoriasis treated with methotrexate [4 developed fibrosis, 4 cirrhosis]; early changes were focal interface hepatitis, followed by entry of fibrous septa, that then linked portal areas, that could lead to micronodular cirrhosis).
McIntosh S, Davidson DL, O'Brien RT, Pearson HA. (1977). Methotrexate hepatotoxicity in children with leukemia. J Pediatr. (8 children treated with methotrexate [1-11 g/m^2^] for leukemia underwent liver biopsy, and 5 had fibrosis; all had at least transient AST elevations [peak 49-400 U/L]).
Ruymann FB, Mosijczuk AD, Sayers RJ. (1977). Hepatoma in a child with methotrexate-induced hepatic fibrosis. JAMA. (11 year old girl with acute leukemia treated with methotrexate for 6 years died of recurrence; found on autopsy to have hepatic steatosis, fibrosis, nodular liver and a small hepatocellular carcinoma).
Chan H, Evans WE, Pratt CB. (1977). Recovery from toxicity with high-dose methotrexate: prognostic factors. Cancer Treat Rep. (Among 65 patients with cancer given high dose methotrexate with leucovorin rescue, 6 had severe toxicity marked by neutropenia and infections and 3 died with multiorgan failure and sepsis with jaundice and ALT elevations).
Horvath E, Saibil FG, Kovacs K, Kerenyi NA, Ross RC. (1978). Fine structural changes in the liver of methotrexate-treated psoriatics. Digestion. (Electron microscopy was done on 55 liver biopsies from 52 patients with psoriasis, 47 on methotrexate therapy; most common findings were diverse mitochondrial abnormalities, detachment of desmosomal plaques and hyperplasia of stellate cells, but these changes did not correlate with duration of therapy or hepatic injury as shown by light microscopy).
Perez C, Sutow WW, Wang YM, Herson J. (1979). Evaluation of overall toxicity of high-dosage methotrexate regimens. Med Pediatr Oncol. (Among 349 courses of high dose methotrexate with leucovorin rescue, AST elevations occurred after 59% with values >3 times ULN in 16%; however, all resolved).
Plomteux G, Closon MT. (1979). Med Chir Dig.
Vaughan WP, Wilcox PM, Alderson PO, Ettinger DS, Abeloff MD. (1979). Hepatic toxicity of adjuvant chemotherapy for carcinoma of the breast. Med Pediatr Oncol. (Four patients being treated with cyclophosphamide, methotrexate and 5-fluouracil developed focal defects on liver scans which were thought to be metastases, but later presumed due to hepatotoxicity with only minor elevations in AST and Alk P, injury being attributed to methotrexate).
Nyfors A. (1980). Methotrexate therapy of psoriasis. Effect and side effects with particular reference to hepatic changes. A survey. Dan Med Bull. (Extensive review of history of development of methotrexate, changes in dosing schedules and evolution of understanding of hepatotoxicity with detailed analysis of liver histology).
Parker D, Bate CM, Craft AW, Graham-Pole J, Malpas JS, Stansfeld AG. (1980). Liver damage in children with acute leukaemia and non-Hodgkin's lymphoma on oral maintenance chemotherapy. Cancer Chemother Pharmacol. (36 children on maintenance chemotherapy for leukemia or lymphoma with methotrexate [25-30 mg/m^2^] and mercaptopurine had frequent AST and Alk P elevations; 8 had liver biopsy which were abnormal in 6 with cirrhosis in 1, no anti-HCV testing available).
Robinson JK, Baughman RD, Auerbach R, Cimis RJ. (1980). Methotrexate hepatotoxicity in psoriasis. Consideration of liver biopsies at regular intervals. Arch Dermatol. (Among 131 liver biopsies done in 43 patients with psoriasis on methotrexate, fibrosis [grade IIIA or B changes] found in 11 after 1-6 years of therapy [total dose 0.6-2.7 g], not predicted by ALT or AST values, but did correlate with older age and total duration of treatment).
Zachariae H, Kragballe K, Søgaard H. (1980). Methotrexate induced liver cirrhosis. Studies including serial liver biopsies during continued treatment. Br J Dermatol. (Analysis of 764 liver biopsies done on 328 patients with psoriasis; 2 had cirrhosis before therapy [0.6%], rising to 13.5% after 2 years and 26% after 5 years; often nonprogressive and patients tolerated continuation of therapy).
Zachariae H, Kragballe K, Thestrup-Pedersen K, Kissmeyer-Nielsen F. (1980). HLA antigens in methotrexate-induced liver cirrhosis. Acta Derm Venereol. (HLA-typing done on 20 patients with psoriasis and methotrexate related cirrhosis was compared to 44 treated patients without cirrhosis and 1291 controls; found a slight increase in HLA-A1+B8 [25% vs 7% vs 15%]).
Willkens RF, Watson MA, Paxson CS. (1980). Low dose pulse methotrexate therapy in rheumatoid arthritis. J Rheumatol. (32 patients with rheumatoid arthritis were treated with methotrexate [7.5-15 mg/week] for 0.3-5 years; 4 had liver biopsies after 2 years of treatment; in those with liver test abnormalities, mild fatty change in 1).
Eschenbach C, Schmitz-Moormann P, Gutjahr P. (1980). Helv Paediatr Acta. (Child with chronic hepatitis B died of hepatocellular carcinoma 5 years after chemotherapy for acute leukemia using methotrexate).
Kamen BA, Nylen PA, Camitta BM, Bertino JR. (1981). Methotrexate accumulation and folate depletion in cells as a possible mechanism of chronic toxicity to the drug. Br J Haematol. (Red cell folate was decreased in 9 of 12 children on methotrexate and in 3 of 5 liver samples from patients on long term methotrexate).
Roenigk HH, Auerbach R, Maibach HI, Weinstein GD. (1982). Methotrexate guidelines - revised. J Am Acad Dermatol. (Expert review of methotrexate and recommendations for use and monitoring; recommended liver biopsy before starting therapy, ALT testing at 3-4 month intervals and repeat liver biopsy after 1.5 g total dose and based upon relative risk, risk factors being alcohol use, previous arsenic exposure, diabetes, obesity, renal impairment and pretreatment liver pathology).
Ashton RE, Millward-Sadler GH, White JE. (1982). Complications in methotrexate treatment of psoriasis with particular reference to liver fibrosis. J Invest Dermatol. (Among 38 patients with psoriasis undergoing liver biopsy before and during methotrexate therapy, 7 [18%] developed fibrosis and 2 [5%] cirrhosis after 16-38 months [1-3.4 g], of whom 3 had moderate alcohol intake).
Lenler-Petersen P, Søgaard H, Thestrup-Pedersen K, Zachariae H. (1982). Galactose tolerance test and methotrexate-induced liver fibrosis and cirrhosis in patients with psoriasis. Acta Derm Venereol. (A total of 151 galactose elimination tests were done on 45 patients with psoriasis and fibrosis undergoing liver biopsies during methotrexate therapy; abnormal results were found in 6% of 46 patients with normal biopsy, 14% of 105 with fibrosis and 20% of 41 with cirrhosis).
Zachariae H, Bjerring P. (1982). Methotrexate in psoriasis with and without leucovorin: effect of different dosage schedules on acute liver toxicity. Acta Derm Venereol. (Comparison of patients with psoriasis given varying regimens of methotrexate [5 mg over 3 days vs 25 mg once weekly, orally vs intramuscularly, with and without leucovorin] found no difference in AST increase during week after dosing [110-187% increase compared to baseline]).
Geronemus RG, Auerbach R, Tobias H. (1982). Liver biopsies upsilon liver scans in methotrexate-treated patients with psoriasis. Arch Dermatol. (Technetium 99m sulfur-colloid scans were not accurate in detecting fibrosis in patients with psoriasis on methotrexate, being abnormal in 6 of 17 patients with normal liver histology and 2 of 5 with fibrosis).
Lawrence CM, Strange RC, Summerly RA, Scriven AJ, Elmahallowy M, Wood A, Fletcher PJ, et al. (1983). Assessment of liver function using fasting bile salt concentrations in psoriasis prior to and during methotrexate therapy. Clin Chim Acta. (Fasting bile acid levels were measured in 18 patients with psoriasis before therapy and 21 receiving long term methotrexate; elevations in bile acids were more accurate than routine liver tests in predicting severe histological abnormalities, but were not sufficiently reliable to detect moderate or severe histological changes).
Beck HI, Foged EK. (1983). Toxic hepatitis due to combination therapy with methotrexate and etretinate in psoriasis. Dermatologica. (47 year old with psoriasis who had been on oral weekly methotrexate for 10 years with normal liver tests, developed fever, jaundice and ascites 4 months after adding 25-75 mg/day etretinate [AST 460 U/L, Alk P 1.5 times ULN, bilirubin 17 mg/dL, prothrombin index 27%], with resolution 2 months after stopping both agents; liver biopsy later showed cirrhosis).
Breithaupt H, Küenzlen E. (1983). High-dose methotrexate for osteosarcoma: toxicity and clinical results. Oncology. (9 patients with osteosarcoma received 122 infusions of high dose methotrexate with leucovorin rescue; "Mild to moderate elevations of serum transaminases have been recorded in nearly each course, usually returning to normal values within 1 week." One patient developed nausea with ALT 1090 U/L and normal bilirubin and with recurrence on re-infusion).
Groff GD, Shenberger KN, Wilke WS, Taylor TH. (1983). Low dose oral methotrexate in rheumatoid arthritis: an uncontrolled trial and review of the literature. Semin Arthritis Rheum. (Retrospective analysis of 28 patients with rheumatoid arthritis treated with methotrexate for 4-30 months; 3 had liver biopsies for elevated serum enzymes and all 3 were normal).
Hoffmeister RT. (1983). Methotrexate therapy in rheumatoid arthritis: 15 years experience. Am J Med. (Retrospective analysis of 78 patients with rheumatoid arthritis treated with methotrexate for up to 15 years; 34 patients underwent 67 liver biopsies, 50 biopsies were normal and 17 showed mild abnormalities with fat and inflammation, 7 with portal fibrosis but none with cirrhosis).
Hilgers RD, Alberts DS, Standefer JC, Skipper BE, Miles NJ, Borst J. (1984). Phase II and pharmacokinetics study of high-dose methotrexate in the treatment of advanced gynecologic malignancy. Gynecol Oncol. (Among 15 patients with gynecological malignancies given several courses of high dose intravenous methotrexate [0.5-8 g/m^2^] with leucovorin rescue, AST elevations occurred during 6% of courses, but all were asymptomatic and resolved).
Haim N, Kedar A, Robinson E. (1984). Methotrexate-related deaths in patients previously treated with cis-diamminedichloride platinum. Cancer Chemother Pharmacol. (6 patients with cancer receiving high dose methotrexate [40 mg/m^2^] and cis-diamminedichloride platinum [CDDP] died with severe stomatitis, fever and leucopenia followed by renal and hepatic failure; the CDDP perhaps causing excessive methotrexate toxicity because of its nephrotoxicity).
Birnie GG, Fitzsimons CP, Czarnecki D, Cooke A, Scobie G, Brodie MJ. (1985). Hepatic metabolic function in patients receiving long-term methotrexate therapy: comparison with topically treated psoriatics, patient controls and cirrhotics. Hepatogastroenterology. (Indocyanine green and antipyrine clearance were measured in 11 patients with psoriasis on long term methotrexate [iv every 2 weeks for 1-16 years] and 14 patients not on therapy and compared to routine liver tests; patients on methotrexate had lower clearances, but there was complete overlap with normal subjects).
Hendel J, Poulsen H, Nyfors B, Nyfors A. (1985). Changes in liver histology during methotrexate therapy of psoriasis correlated to the concentration of methotrexate and folate in erythrocytes. Acta Pharmacol Toxicol (Copenh). (Among 31 patients with psoriasis on methotrexate therapy, liver biopsies showed mild to moderate fatty change and none had progression of fibrosis, but abnormalities that did occur correlated with lower red cell folate and higher methotrexate levels).
Weinblatt ME, Coblyn JS, Fox DA, Fraser PA, Holdsworth DE, Glass DN, Trentham DE. (1985). Efficacy of low dose methotrexate in rheumatoid arthritis. N Engl J Med. (Placebo controlled crossover trial of methotrexate [7.5-15 mg/week] for 24 weeks in 33 patients with severe rheumatoid arthritis; abnormal ALT or AST occurred in 21% on drug and 3% on placebo, all episodes resolving rapidly with holding the dose).
van de Kerkhof PC, Hoefnagels WH, van Haelst UJ, Mali JW. (1985). Methotrexate maintenance therapy and liver damage in psoriasis. Clin Exp Dermatol. (Among 44 patients with psoriasis treated with methotrexate for 3 to 15 years, 7 [16%] had fibrosis and 2 [4.5%] cirrhosis, no correlation with ALT or AST elevations and poor correlation with total dose; more common in elderly; all received >2 g total dose).
Williams HJ, Willkens RF, Samuelson CO, Alarcon GS, Guttadauria M, Yarboro C, Polisson RP, et al. (1985). Comparison of low-dose oral pulse methotrexate and placebo in the treatment of rheumatoid arthritis: a controlled clinical trial. Arthritis Rheum. (Controlled trial of methotrexate [7.5-15 mg/week] vs placebo for 18 weeks in 189 patients with rheumatoid arthritis; ALT elevations >2 times ULN occurred in 19% of 95 patients on methotrexate vs 3% of 94 on placebo; most common cause of drug withdrawal).
Lanse SB, Arnold GL, Gowans JD, Kaplan MM. (1985). Low incidence of hepatotoxicity associated with long-term, low-dose oral methotrexate in treatment of refractory psoriasis, psoriatic arthritis, and rheumatoid arthritis. An acceptable risk/benefit ratio. Dig Dis Sci. (Serial liver biopsies among 30 patients with psoriasis or rheumatoid arthritis treated with oral methotrexate weekly showed normal results in 50% and all remained normal on repeat biopsy 1-10 years later; among 11 with fat and 4 with mild fibrosis initially, 4 worsened, 8 were unchanged and 3 were better in follow up and none developed cirrhosis).
Mackenzie AH. (1985). Hepatotoxicity of prolonged methotrexate therapy for rheumatoid arthritis. Cleve Clin Q. (Among 60 patients with rheumatoid arthritis being treated with methotrexate who underwent liver biopsy, none had fibrosis; and rates of steatosis [50% vs 44%] and portal inflammation [18% vs 20%] were not increased compared to controls).
Pestana A, Halprin KM, Taylor JR, Schiff ER, Esquenazi V, Comerford M, Gomez C. (1985). Predictive value of HLA antigen for methotrexate-induced liver damage in patients with psoriasis. J Am Acad Dermatol. (Among 32 patients with psoriasis treated with methotrexate for at least 4 years who had variable degrees of hepatic fibrosis, HLA typing showed no association with degree of fibrosis or cirrhosis).
Tolman KG, Clegg DO, Lee RG, Ward JR. (1985). Methotrexate and the liver. J Rheumatol Suppl. (Analysis of liver biopsies in 29 patients with rheumatoid arthritis on weekly methotrexate for at least 2 years, found 24% normal, 41% with mild changes, 34% with fibrosis and none with cirrhosis; ALT levels did not predict more severe histologic changes; hypoalbuminemia and persistent ALT elevations were somewhat predictive and significant abnormalities found only after 1.5 g total dose).
Weinstein A, Marlowe S, Korn J, Farouhar F. (1985). Low-dose methotrexate treatment of rheumatoid arthritis. Long-term observations. Am J Med. (Among 25 patients with rheumatoid arthritis treated with methotrexate for 0.5 to 5 years, ALT elevations found in 48% at least once; 6 of 17 [35%] had fibrosis on liver biopsy but none had cirrhosis; histology having a poor correlation with ALT elevations).
Miller JA, Dodd H, Rustin MHA, Lees WR, Levene GM, Kirby JD, Munro DD. (1985). Ultrasound as a screening procedure for methotrexate-induced hepatic damage in severe psoriasis. Br J Dermatol. (Among 82 patients with psoriasis on methotrexate, abnormal ultrasound findings [moderate-severe fat or fibrosis] found in 22% of those with normal [n=49], 73% of those with abnormal liver biopsies without fibrosis [n=30] and all with fibrosis [n=8]).
Jones SK, Aherne GW, Campbell MJ, White JE. (1986). Methotrexate pharmacokinetics in psoriatic patients developing hepatic fibrosis. Arch Dermatol. (Pharmacokinetic studies on 7 patients with psoriasis with fibrosis due to methotrexate and 12 without fibrosis showed no differences in peak levels of methotrexate or rates of clearance).
Kremer JM, Lee JK. (1986). The safety and efficacy of the use of methotrexate in long-term therapy for rheumatoid arthritis. Arthritis Rheum. (Among 29 patients with rheumatoid arthritis treated with methotrexate for 7-54 months, 69% had at least one AST elevation, occurring randomly and not requiring dose change; comparison of 29 baseline and 31 follow up liver biopsies showed minimal worsening and no correlation with AST elevations).
Kremer JM, Galivan J, Streckfuss A, Kamen B. (1986). Methotrexate metabolism analysis in blood and liver of rheumatoid arthritis patients: association with hepatic folate deficiency and formation of polyglutamates. Arthritis Rheum. (Among 29 patients with rheumatoid arthritis, measurement of folate metabolites in liver tissue showed evidence of folate deficiency in all patients on methotrexate which was restored by oral folate therapy).
Reynolds FS, Lee WM. (1986). Hepatotoxicity after long-term methotrexate therapy. South Med J. (Among 14 patients with psoriasis who underwent liver biopsy, 4 [27%] had fibrosis all of whom had been treated for more than 5 years).
Berkowitz RS, Goldstein DP, Bernstein MR. (1986). Ten years' experience with methotrexate and folinic acid as primary therapy for gestational trophoblastic disease. Gynecol Oncol. (Among 185 patients with gestational trophoblastic disease treated with methotrexate and leucovorin rescue, sustained remission in 82% with one course; hepatotoxicity occurred in 14% but abnormalities returned to normal within 2 weeks).
Rademaker M, Webb JA, Lowe DG, Meyrick-Thomas RH, Kirby JD, Munro DD. (1987). Magnetic resonance imaging as a screening procedure for methotrexate induced liver damage. Br J Dermatol. (Among 51 patients with psoriasis on methotrexate therapy, magnetic resonance imaging liver parameters did not correlate with either steatosis or fibrosis on liver biopsy).
Gispen JG, Alarcón GS, Johnson JJ, Acton RT, Barger BO, Koopman WJ. (1987). Toxicity of methotrexate in rheumatoid arthritis. J Rheumatol. (Among 72 patients with rheumatoid arthritis treated with oral methotrexate weekly, 55% had benefit and 74% had side effects, usually minor, but 7 were serious and 2 patients died both related to leukopenia and infection and not to liver injury).
Leonard PA, Clegg DO, Carson CC, Cannon GW, Egger MJ, Ward JR. (1987). Low dose pulse methotrexate in rheumatoid arthritis: an 8-year experience with hepatotoxicity. Clin Rheumatol. (Among 163 patients with rheumatoid arthritis treated with methotrexate for 0.3-7 years [total dose 0.1-3.1 g], serum enzyme elevations occurred at least once in 58% but led to discontinuation in only 5%; elevations did not correlate with alcohol use, age, dose or days relative to methotrexate dose).
Williams CN, McCauley D, Malatjalian DO, Turnbull GK, Ross JB. (1987). The aminopyrine breath test, an inadequate early indicator of methotrexate-induced liver disease in patients with psoriasis. Clin Invest Med. (Among 32 patients with psoriasis on methotrexate therapy, aminopyrine breath tests were abnormal [<7%] in none of 24 without fibrosis and 3 of 8 with fibrosis and, thus, were not accurate enough to replace liver biopsy in assessing progressive injury).
Shepard KV, Levin B, Faintuch J, Doria MI, DuBrow RA, Riddell RH. (1987). Hepatitis in patients receiving intraarterial chemotherapy for metastatic colorectal carcinoma. Am J Clin Oncol. (Among 51 patients with metastatic colon cancer treated with hepatic intra-arterial floxuridine [FUDR] and dichloromethotrexate or mitomycin, 47% developed liver injury and 25% were jaundiced, usually within 1-8 weeks of the first cycle [ALT 26-710 U/L, bilirubin 3-12.5 mg/dL], resolving in 1 week to 3 months, but two developed biliary stricture, cause likely to be FUDR).
Fried M, Kalra J, Ilardi CF, Sawitsky A. (1987). Hepatocellular carcinoma in a long-term survivor of acute lymphocytic leukemia. Cancer. (28 year old woman presented with hepatocellular carcinoma and cirrhosis 22 years after diagnosis of acute leukemia treated successfully with mercaptopurine and methotrexate [6 years: total dose 4 g], with ALT 90 U/L, Alk P 538 U/L, bilirubin 1.3 mg/dL; no other cause of cirrhosis found, but published before availability of tests for hepatitis C).
Szanto E, Sandstedt B, Kollberg B. (1987). Hepatotoxicity associated with low-dose, long-term methotrexate treatment of rheumatoid arthritis. Scand J Rheumatol. (Among 17 patients with rheumatoid arthritis treated with methotrexate for 1-5 years, liver biopsies were normal in 16 with only mild fatty change and nuclear variability; 1 patient had mild fibrosis [0.6 g total dose and normal ALT levels]).
Weber BL, Tanyer G, Poplack DG, Reaman GH, Feusner JH, Miser JS, Bleyer WA. (1987). Transient acute hepatotoxicity of high-dose methotrexate therapy during childhood. NCI Monogr. (Among 24 children with acute leukemia treated with 75 cycles of very high dose methotrexate [33.6 g/24 hr] and leucovorin rescue, ALT elevations occurred in 30% after first course but in >92% after 3 courses, values reaching 1500 U/L, Alk P and bilirubin elevations peaking later, sometimes with symptoms, but without any long term clinically apparent consequences).
Zachariae H, Schrøder H, Foged E, Søgaard H. (1987). Methotrexate hepatotoxicity and concentrations of methotrexate and folate in erythrocytes - relation to liver fibrosis and cirrhosis. Acta Derm Venereol. (Assessment of red cell folate levels and liver histology in 30 patients with psoriasis receiving long term methotrexate therapy found no correlation of folate levels with severity of liver injury, duration of therapy or dose).
Zachariae H, Søgaard H. (1987). Methotrexate-induced liver cirrhosis. A follow-up. Dermatologica. (Analysis of 113 liver biopsies from 25 patients with psoriasis who developed cirrhosis on methotrexate therapy; cirrhosis found after 0.6-10 g [mean=3.1 g] of methotrexate; 21 patients were continued on therapy [at lowest possible dose and with prohibition against alcohol] for up to 9 years without evidence of worsening liver disease or clinical decompensation).
Hendel J, Poulsen H, Nyfors B, Nyfors A. (1985). Changes in liver histology during methotrexate therapy of psoriasis correlated to the concentration of methotrexate and folate in erythrocytes. Acta Pharmacol Toxicol (Copenh). (Letter in response to Zachariae et al. [1987] stressing the need to monitor serial red blood cell folate levels in assessing methotrexate hepatotoxicity).
Aponte J, Petrelli M. (1988). Histopathologic findings in the liver of rheumatoid arthritis patients treated with long-term bolus methotrexate. Arthritis Rheum. (Among 23 patients with rheumatoid arthritis treated with methotrexate for more than 1 years [total dose 4.7-10.2 g] using weekly regimens, 52% had serum enzyme elevations and 21 underwent liver biopsy which was normal in 68% and showed mild fibrosis in 24%; none had severe fibrosis or cirrhosis).
Paramsothy J, Strange R, Shariff H, Collins M, Shaw P, Lawrence CM. (1988). The use of antipyrine clearance to measure liver damage in patients receiving methotrexate. Br J Dermatol. (Among 15 patients with psoriasis on methotrexate, antipyrine saliva clearance tests correlated with degree of liver abnormality, but without clear demarcation of abnormal result).
Banerjee AK, Lakhani S, Vincent M, Selby P. (1988). Dose-dependent acute hepatitis associated with administration of high dose methotrexate. Hum Toxicol. (18 year old girl with osteosarcoma given high dose methotrexate [20 g] and leucovorin rescue had rise of ALT to 908 U/L at day 10, rapidly falling to normal with minimal rise with subsequent dose of 0.8 g intravenously).
Bjorkman DJ, Hammond EH, Lee RG, Clegg DO, Tolman KG. (1988). Hepatic ultrastructure after methotrexate therapy for rheumatoid arthritis. Arthritis Rheum. (Liver biopsy analyses in 26 patients treated with methotrexate for 1 to 10 years, most had some abnormality and all had increased collagen in space of Disse by electron microscopy; by light microscopy, 62% had steatosis, 12% inflammation and 15% mild pericentral fibrosis not seen in control biopsy material).
Kevat S, Ahern M, Hall P. (1988). Hepatotoxicity of methotrexate in rheumatic diseases. Med Toxicol Adverse Drug Exp. (Detailed review of liver histology changes associated with methotrexate use and authors' recommendations for liver biopsy before and during therapy [after 1.5 g and every 2 years thereafter]).
Lewis JH, Schiff E. (1988). Methotrexate-induced chronic liver injury: guidelines for detection and prevention. The ACG Committee on FDA-related matters. American College of Gastroenterology. Am J Gastroenterol. (Review of methotrexate induced liver disease and recommendations for monitoring).
Kremer JM, Lee JK. (1988). A long-term prospective study of the use of methotrexate in rheumatoid arthritis. Update after a mean of fifty-three months. Arthritis Rheum. (Further follow up on cohort of 29 patients with rheumatoid arthritis treated with methotrexate for average of 4 years [2.5-6 years] found sustained improvements in 25 patients, 22 had at least one elevation in AST levels).
Risteli J, Sød H, Oikarinen A, Risteli L, Karvonen J, Zachariae H. (1988). Aminoterminal propeptide of type III procollagen in methotrexate-induced liver fibrosis and cirrhosis. Br J Dermatol. (Among 24 patients with psoriasis on methotrexate therapy, PIIIP elevations found in none of 9 with normal liver biopsy, 5 of 9 with fibrosis and 2 of 5 with cirrhosis).
Shergy WJ, Polisson RP, Caldwell DS, Rice JR, Pisetsky DS, Allen NB. (1988). Methotrexate-associated hepatotoxicity: retrospective analysis of 210 patients with rheumatoid arthritis. Am J Med. (Analysis of 538 liver biopsies done on 399 patients with various diagnoses being monitored during methotrexate therapy, found 2 with cirrhosis and 12 with fibrosis; but only 6 of 210 patients with rheumatoid arthritis had fibrosis and none had cirrhosis; the 6 with fibrosis included 5 with obesity, 3 with diabetes, but only one with liver test abnormalities [all <2 times ULN]).
Weinblatt ME, Trentham DE, Fraser PA, Holdsworth DE, Falchuk KR, Weissman BN, Coblyn JS. (1988). Long-term prospective trial of low-dose methotrexate in rheumatoid arthritis. Arthritis Rheum. (Among 26 patients with rheumatoid arthritis treated long term, 8 [31%] had ALT or AST elevations >2 times ULN, but all resolved and none required permanent discontinuation; liver biopsies done in 17 showed no fibrosis, but minor degrees of fat and inflammation [15 grade I, 2 grade II Roenigk changes]).
Roenigk HH, Auerbach R, Maibach HI, Weinstein GD. (1988). Methotrexate in psoriasis: revised guidelines. J Am Acad Dermatol. (Expert advice and guidelines for use of methotrexate in psoriasis; recommends pretreatment liver biopsy, serum enzymes every 3-4 months, biopsy after 1.5 g total dose and repeat biopsies based upon liver test abnormalities and second biopsy results; discusses Roenigk grading system of I-IV and recommends stopping methotrexate if grades IIIB or IV are found).
Alarcón GS, Tracy IC, Blackburn WD. (1989). Methotrexate in rheumatoid arthritis. Toxic effects as the major factor in limiting long-term treatment. Arthritis Rheum. (Among 152 patients with rheumatoid arthritis started on methotrexate, only 50% remained on long-term [>5 year] therapy; toxicity accounted for 60% of discontinuations; none were hepatic and liver biopsies in 9 showed no fibrosis).
McKendry RJ, Cyr M. (1989). Toxicity of methotrexate compared with azathioprine in the treatment of rheumatoid arthritis. A case-control study of 131 patients. Arch Intern Med. (Among 131 patients with rheumatoid arthritis treated for up to 5 years, elevated liver tests > twice the ULN occurred in 14% of 94 patients on methotrexate vs none of 37 on azathioprine).
Bridges SL, Alarcón GS, Koopman WJ. (1989). Methotrexate-induced liver abnormalities in rheumatoid arthritis. J Rheumatol. (Editorial on hepatotoxicity of methotrexate in rheumatoid arthritis comments on the infrequency of significant fibrosis in cohorts studied from the United States and recommends that routine pretreatment and during-treatment liver biopsies are not needed in patients with normal liver tests and no risk factors for liver disease).
Clegg DO, Furst DE, Tolman KG, Pogue R. (1989). Acute, reversible hepatic failure associated with methotrexate treatment of rheumatoid arthritis. J Rheumatol. (Two women with rheumatoid arthritis developed liver disease on methotrexate; 38 year old developed steatosis and fibrosis after 4 years and cirrhosis with ascites after 5 years, improving on stopping therapy: Case 1; 54 year old with mild fibrosis on liver biopsy before therapy developed ascites and jaundice after two years, improving on stopping methotrexate).
O'Connor GT, Olmstead EM, Zug K, Baughman RD, Beck JR, Dunn JL, Seal P, et al. (1989). Detection of hepatotoxicity associated with methotrexate therapy for psoriasis. Arch Dermatol. (Retrospective analysis of 147 liver biopsies done in 78 patients with psoriasis treated with methotrexate found fibrosis or cirrhosis in 5 [10%] before and 23 [24%] on therapy; individual liver tests had poor sensitivity and specificity for detecting fibrosis, but authors developed an algorithm with reasonable accuracy; final model included age, sex, AST, Alk P, cholecystitis history and cumulative dose).
Kremer JM, Lee RG, Tolman KG. (1989). Liver histology in rheumatoid arthritis patients receiving long-term methotrexate therapy: a prospective study with baseline and sequential biopsy samples. Arthritis Rheum. (27 patients with rheumatoid arthritis treated with methotrexate for 1-6 years underwent 101 liver biopsies; no patient had fibrosis on pretreatment biopsy, but rates increased to 8% at 2, 16% at 3, and 40% at 4 years; correlated with duration of therapy, patient age and history of alcohol use, but not AST or ALT elevations which were often raised; no cirrhosis).
Kremer JM, Kaye GI. (1989). Electron microscopic analysis of sequential liver biopsy samples from patients with rheumatoid arthritis: correlation with light microscopic findings. Arthritis Rheum. (Analysis of 52 liver biopsies from 22 patients with rheumatoid arthritis treated with methotrexate for 2-6 years found only minor, nonspecific changes by electron microscopy).
Rau R, Karger T, Herbern G, Fernzel H. (1989). Liver biopsy findings in patients with rheumatoid arthritis undergoing long-term treatment with methotrexate. J Rheumatol. (Analysis of liver biopsies from 60 patients with rheumatoid arthritis, comparing 60 from before therapy to 40 taken during therapy [mean total dose 1.3 g] found no significant difference using a semiquantitative analysis of 10 features including fibrosis, fat, ballooning, necrosis and inflammation; normal findings in 68% before vs 58% on therapy, fibrosis in 15% vs 25%; ALT elevations in 15% vs 50%).
Newman M, Auerbach R, Feiner H, Holzman RS, Shupack J, Migdal P, Culubret M, et al. (1989). The role of liver biopsies in psoriatic patients receiving long-term methotrexate treatment improvement in the abnormalities after cessation of treatment. Arch Dermatol. (Retrospective analysis of 364 liver biopsies from 168 patients with psoriasis treated with methotrexate for 0 to 19 years [mean=4 years]; among 83 biopsies before therapy, 80% were normal, 20% had fibrosis, none cirrhosis [those with cirrhosis were not treated]; during treatment, fibrosis scores increased but rarely by much and most improved with subsequent withdrawal of therapy).
Brick JE, Moreland LW, Al-Kawas F, Chang WWL, Layne RD, DiBartolomeo AG. (1989). Prospective analysis of liver biopsies before and after methotrexate therapy in rheumatoid arthritis patients. Semin Arthritis Rheum. (Among liver biopsies done in 96 patients with rheumatoid arthritis before or after methotrexate therapy, fibrosis was found in 3% of 62 pretreatment and 10-12% of 88 posttreatment biopsies, cirrhosis was found in 2 patients, but alcohol was blamed in one instance).
Zachariae H, Søgaard H, Heickendorff L. (1989). Serum aminoterminal propeptide of type III procollagen. A non-invasive test for liver fibrogenesis in methotrexate-treated psoriatics. Acta Derm Venereol. (Serum PIIIP levels were assessed in 72 patients with psoriasis before or during methotrexate therapy; mean levels were higher in patients with fibrosis [5.2 vs 3.3 µg/L] but considerable overlap in values; serial results in 11 patients were normal in most).
Drosos AA, Psychos D, Andonopoulos AP, Stefanaki-Nikou S, Tsianos EB, Moutsopoulos HM. (1990). Methotrexate therapy in rheumatoid arthritis. A two year prospective follow-up. Clin Rheumatol. (Among 130 Greek patients with rheumatoid arthritis treated with methotrexate [7.5-15 mg/week] for up to 2 years, 25% developed raised serum enzymes, requiring discontinuation in 4%; liver biopsies in 41 patients [mean total dose 1550 mg] showed mild fibrosis in 15%, no cirrhosis and no correlation with ALT elevations).
Fries JF, Singh G, Lenert L, Furst DE. (1990). Aspirin, hydroxychloroquine, and hepatic enzyme abnormalities with methotrexate in rheumatoid arthritis. Arthritis Rheum. (Among "nearly" 2,600 patients with rheumatoid arthritis in the ARAMIS database, abnormal ALT values were present in <5%, highest rates in those on salicylates [7.6%], sulindac [8.3%], methotrexate [9.5%] and lowest in those on hydroxychloroquine even in combination with methotrexate and salicylates).
Flowers MA, Heathcote J, Wanless IR, Sherman M, Reynolds WJ, Cameron RG, Levy GA, et al. (1990). Fulminant hepatitis as a consequence of reactivation of hepatitis B virus infection after discontinuation of low-dose methotrexate therapy. Ann Intern Med. (57 year old woman with rheumatoid arthritis and inactive HBsAg carrier state, developed severe hepatitis 22 days after stopping methotrexate [given for 7 years] for pulmonary toxicity with appearance of HBV DNA and IgM anti-HBc, progression to hepatic failure and successful liver transplantation after which she remained HBsAg positive; use of corticosteroids not mentioned).
Gilbert SC, Klintmalm G, Menter A, Silverman A. (1990). Methotrexate-induced cirrhosis requiring liver transplantation in three patients with psoriasis. A word of caution in light of the expanding use of this 'steroid-sparing' agent. Arch Intern Med. (Three patients with psoriasis underwent liver transplantation for methotrexate induced cirrhosis; ages 39, 46 and 59 years, treated for 5, 10 and 12 years, total doses of 9.5-26 g, presenting with anasarca, liver failure and variceal hemorrhage, two survived and had excellent remission in psoriasis; none had undergone surveillance liver biopsies; no mention of hepatitis C testing or alcohol history).
Kaito K, Katayama T, Yoshida M, Saito A, Kobayashi M, Ochiai S, Masuoka S, et al. (1990). Rinsho Ketsueki.
Keim D, Ragsdale C, Heidelberger K, Sullivan D. (1990). Hepatic fibrosis with the use of methotrexate for juvenile rheumatoid arthritis. J Rheumatol. (17 year old girl with juvenile rheumatoid arthritis had a normal liver biopsy after 1.5 years of methotrexate therapy, but had mild fibrosis (Roenigk IIIA) on biopsy after 3.5 years and methotrexate was stopped; AST levels were minimally and transiently elevated during the first 2 years of therapy and repeatedly normal thereafter).
Gabriel S, Cregsen E, O'Fallen WM, Jaquith J, Bunch T. (1990). Treatment of rheumatoid arthritis with higher dose intravenous methotrexate. J Rheumatol. (Pilot study of intravenous, higher dose methotrexate for resistant rheumatoid arthritis; AST values increased by an average of 13 U/L; maximum level was 50 U/L).
Furst DE, Erickson N, Clute L, Koehnke R, Burmeister L, Kohler J. (1990). Adverse experience with methotrexate during 176 weeks of a long-term prospective trial in rheumatoid arthritis patients. J Rheumatol. (Among 45 patients with rheumatoid arthritis treated with methotrexate for up to 3 years, 97% had side effects leading to dose modifications in 71%; ALT elevations above 3 times ULN occurred in 33% of patients, but were usually not a reason for changing the dose on their own).
Mitchell D, Smith A, Rowan B, Warnes TW, Haboubi NY, Lucas SB, Chalmers RJ. (1990). Serum type III procollagen peptide, dynamic liver function tests and hepatic fibrosis in psoriatic patients receiving methotrexate. Br J Dermatol. (PIIIP levels were measured in 51 patients with psoriasis on methotrexate for 1-13 years [10 with fibrosis, 3 cirrhosis] and controls; levels were often raised in treated patients [69%], but with somewhat poor correlation to hepatic histology and serum enzyme elevations; BSP and galactose clearance tests were similarly poorly predictive and of limited practicality).
Willkens RF, Leonard PA, Clegg DO, Tolman KG, Ward JR, Marks CR, Greene ML, et al. (1990). Liver histology in patients receiving low dose pulse methotrexate for the treatment of rheumatoid arthritis. Ann Rheum Dis. (Liver biopsies were done on 52 patients with rheumatoid arthritis treated with methotrexate [7.5-15 mg/week] for 2-8 years [773-3913 mg]; fibrosis found in 29%, cirrhosis in none, and only 2 were normal; grade of abnormality did not correlate with age, duration of treatment, total dose or serum enzyme elevations [elevated at least once in 90%]).
Odeh M. (1990). Methotrexate, liver abnormalities and RA. J Rheumatol. (Letter in response to Rau et al. [1989] arguing against the conclusion that methotrexate does not induce liver injury; reply by the authors).
Kujala GA, Shamma'a JM, Chang WL, Brick JE. (1990). Hepatitis with bridging fibrosis and reversible hepatic insufficiency in a woman with rheumatoid arthritis taking methotrexate. Arthritis Rheum. (58 year old woman with rheumatoid arthritis on oral methotrexate 10 mg weekly for 6 years [2.7 g total dose] developed ascites with bilirubin 1.6 mg/dL, Alk P 100 U/L, ALT 12 U/L, albumin 3 g/dL, platelets 133,000 μ/L, liver biopsy showing bridging fibrosis, responding to diuretics).
Zachariae H. (1990). Methotrexate side-effects. Br J Dermatol. (Review of side effects of methotrexate; table showing results of 25 patients with psoriasis who developed cirrhosis after 1-10 years of therapy [total dose 0.5-6.5 g], many of whom were able to continue methotrexate for another 1-8 years).
Weinblatt ME, Kaplan H, Germain BF, Merriman RC, Solomon SD, Wall B, Anderson L, et al. (1990). Low-dose methotrexate compared with auranofin in adult rheumatoid arthritis. A thirty-six-week, double-blind trial. Arthritis Rheum. (Among 281 patients with rheumatoid arthritis treated for 36 weeks, those treated with methotrexate had higher, earlier and better clinical responses; ALT elevations >2 times ULN occurred in 24% of methotrexate- vs 7% of gold-treated patients, requiring discontinuation in 6% vs 1.4%).
Schmiegelow K, Pulczynska M. (1990). Prognostic significance of hepatotoxicity during maintenance chemotherapy of childhood acute leukemia. Br J Cancer. (Among 115 children on maintenance chemotherapy for leukemia with methotrexate and mercaptopurine, ALT levels were on average elevated [>40 U/L] in 60% and this group had a lower rate of relapse; elevations tended to decrease over time during long-term therapy).
Rose CD, Singsen B, Eichenfield AH, Goldsmith DP, Athreya BH. (1990). Safety and efficacy of methotrexate therapy for juvenile rheumatoid arthritis. J Pediatr. (29 children with juvenile rheumatoid arthritis were treated with methotrexate [~7 mg/m^2^/week] for 8 to 39 months; >80% response rate and only 1 child had ALT elevations, which were transient, resolving with dose reduction).
Martini A, Ravelli A, Viola S, Burgio RG. (1991). Methotrexate hepatotoxic effects in children with juvenile rheumatoid arthritis. J Pediatr. (Letter in response to Rose et al. [1990]; authors treated 27 children with methotrexate for 6 to 30 months [~9 mg/m^2^] with 74% response rate; 56% had ALT elevations, all self-limiting or resolving with stopping).
Zachariae H, Aslam HM, Bjerring P, Sogaard H, Zachariae E, Heickendorff L. (1991). Serum aminoterminal propeptide of type III precollagen in psoriasis and psoriatic arthritis: relation to liver fibrosis and arthritis. J Am Acad Dermatol. (PIIIP levels were assessed in 170 patients with psoriasis being treated with methotrexate; levels were usually elevated in those with psoriatic arthritis [38% without fibrosis], but elevations in those with psoriasis alone were reliable markers for fibrosis or cirrhosis on liver biopsy [67% of 24] vs nonspecific or normal findings [4% of 52]; no correlation between ALT and PIIIP levels).
Mehdi A, Marteau P, Lavergne A, Molho-Sabatier P, Cochand-Priollet B, Caen J, Rambaud JC. (1991). Gastroenterol Clin Biol. (64 year old man with psoriasis presented with 16 cm hepatocellular carcinoma having a history of 2 years of therapy with methotrexate [total dose 3 g] and arsenic [1.5 g] 20 years earlier; negative for HCV, HBV and iron markers).
Scully CJ, Anderson CJ, Cannon GW. (1991). Long-term methotrexate therapy for rheumatoid arthritis. Semin Arthritis Rheum. (Analysis of 124 patients with rheumatoid arthritis treated with methotrexate, 39 for more than 5 years; elevated serum enzymes in 70% which resulted in stopping in 7%; 57 liver biopsies done in 40 patients after mean of 2.7 years [1.3 g] of which 17 [30%] showed fibrosis but none cirrhosis, but only 2 of these stopped therapy).
Hall PD, Ahern MJ, Jarvis LR, Stoll P, Jenner MA, Harley H. (1991). Two methods of assessment of methotrexate hepatotoxicity in patients with rheumatoid arthritis. Ann Rheum Dis. (Comparison of two methods of assessing collagen in serial liver biopsies from 18 patients with rheumatoid arthritis on methotrexate for 1-12 years; mild increases in pericellular collagen were best shown by computerized morphometry, but presence of collagen did not correlate with total methotrexate dose).
Ahern MJ, Kevat S, Hill W, Hayball PJ, Harley H, Hall PD. (1991). Hepatic methotrexate content and progression of hepatic fibrosis: preliminary findings. Ann Rheum Dis. (Among 16 patients with rheumatoid arthritis treated with methotrexate for 1-6 years undergoing paired liver biopsies and quantitative assessment of fibrosis [image analysis], the 3 patients with the most progression [>3.5%] had high levels of methotrexate and its glutamates in liver).
Wolfe F, Cathey MA. (1991). The effect of age on methotrexate efficacy and toxicity. J Rheumatol. (Among 235 patients with rheumatoid arthritis treated with methotrexate, at least one AST elevation occurred in 26% of 51 elderly [>65 years] compared to 31% of 184 younger patients).
Whiting-O'Keefe QE, Fye KH, Sack KD. (1991). Methotrexate and histologic hepatic abnormalities: a meta-analysis. Am J Med. (Metaanalysis of 15 studies of liver histology during long term, low dose methotrexate therapy in psoriasis [n=299] and rheumatoid arthritis [n=334]; progression in one Roenigk score after each gram of methotrexate in 6.9% of patients, correlating with cumulative dose and alcohol use; advanced fibrosis [Roenigk IIIB and IV] in 5%, higher in alcoholics and in psoriasis).
Singh G, Fries JF, Williams CA, Zatarain E, Spitz P, Bloch DA. (1991). Toxicity profiles of disease modifying antirheumatic drugs in rheumatoid arthritis. J Rheumatol. (Analysis of side effects of 7 agents from the ARAMIS database including 2,479 patients with rheumatoid arthritis [497 on methotrexate for 735 person-years] reported 41 instances of liver abnormalities and 2 of jaundice in patients on methotrexate, rates higher than gold, hydroxychloroquine, penicillamine, azathioprine and cyclophosphamide).
Watson RG, Smallwood RA. (1991). Low-dose methotrexate therapy and hepatotoxicity. The view of the hepatologist. Med J Aust. (Editorial on hepatotoxicity of long term, low dose methotrexate therapy stressed the lack of progression of fibrosis found in many publications and that 0-22% of patients had fibrosis and 0-1.5% had cirrhosis even before therapy; "the balance of evidence indicates that the risk of liver damage is small").
Grosflam J, Weinblatt ME. (1991). Methotrexate: mechanism of action, pharmacokinetics, clinical indications, and toxicity. Curr Opin Rheumatol. (Review of recent literature on mechanism of action, pharmacokinetics, clinical indications and toxicity; summary of 7 papers on hepatotoxicity).
Korman MG. (1992). Low-dose methotrexate therapy and hepatotoxicity. Med J Aust. (Letter in response to Watson and Smallwood [1991] questioning wisdom of using routine liver tests to monitor for methotrexate liver injury).
Aponte J, Petrelli M, von Dawson N. (1992). Liver enzyme levels in arthritis patients treated with long-term bolus methotrexate. Arthritis Rheum. (Analysis of ALT, AST and GGT levels in 40 patients treated with methotrexate for more than 10 years found no difference in serum enzymes or liver histology in patients with or without concurrent hydroxychloroquine treatment).
Kremer JM, Phelps CT. (1992). Long term prospective study of the use of methotrexate in the treatment of rheumatoid arthritis: update after mean of 90 months. Arthritis Rheum. (Update on clinical trial of long term methotrexate in 29 patients with rheumatoid arthritis, including 18 patients still on therapy [for 6-9 years; total dose ~6 g]; no discussion of hepatotoxicity).
Kremer JM. (1992). Liver biopsies in patients with rheumatoid arthritis receiving methotrexate. Where are we going?. J Rheumatol. (Editorial on liver biopsy recommendations for patients with rheumatoid arthritis receiving methotrexate; recommended baseline biopsy only for patients with abnormal liver tests or at high risk for having liver disease and repeat biopsy on therapy for repeated AST elevations or decrease in serum albumin, stopping therapy if significant fibrosis is found [Roenigk grade IIIB or IV]).
Tishler M, Caspi D, Halperin Z, Baratz M, Moshkowitz M, Yaron M. (1992). A prospective analysis of liver biopsies in rheumatoid arthritis patients receiving long term methotrexate therapy. Rheumatol Int. (Analysis of paired liver biopsies from 10 patients with rheumatoid arthritis before and after methotrexate therapy for 4-7.5 years [total dose 1.4 to 7.5 g], showed no progression in fibrosis, despite AST elevations in 30%; 1 patient had mild fibrosis before therapy and amount did not change).
Graham LD, Myones BL, Rivas-Chacon RF, Pachman LM. (1992). Morbidity associated with long-term methotrexate therapy in juvenile rheumatoid arthritis. J Pediatr. (Among 62 children with juvenile rheumatoid arthritis treated with methotrexate for 1-6 years, 9 had ALT elevations [119-1500 U/L], resolving with stopping but no recurrence on restarting; liver biopsy in 12 [after 0.8 to 1.4 g] found none with fibrosis).
Locasciulli A, Mura R, Fraschini D, Gornati GL, Scoven E, Gervasoni A, Uderzo C, et al. (1992). High-dose methotrexate administration and acute liver damage in children treated for acute lymphoblastic leukemia. A prospective study. Haematologica. (Among 68 children with acute leukemia treated with high dose methotrexate monitored with liver tests before and 1 and 2 weeks after each of 272 courses, 88% had ALT elevations during induction courses and 38% during consolidation; 85% had mild indirect hyperbilirubinemia, but only 1 patient had hepatotoxicity [peak ALT 700 U/L and jaundice], which resolved rapidly).
Phillips CA, Cera PJ, Mangan TF, Newman ED. (1992). Clinical liver disease in patients with rheumatoid arthritis taking methotrexate. J Rheumatol. (Among 134 patients with rheumatoid arthritis treated with methotrexate, 3 [2%] developed histologic signs of severe liver disease; ages 58-68 years, treated for 2-4 years [total dose 1.3-1.6 g] with biopsy showing advanced fibrosis [n=2] or cirrhosis [n=1], 2 with ascites, 1 died; none were alcoholic, 2 had normal pretreatment biopsy; AST levels elevated on therapy in 2, GGT in the third).
Themido R, Loureiro M, Pecegueiro M, Brandão M, Campos MC. (1992). Methotrexate hepatotoxicity in psoriatic patients submitted to long-term therapy. Acta Derm Venereol. (Analysis of paired liver biopsies done in 30 Portuguese patients with psoriasis before and on methotrexate [0.2-7 g], 8 had fibrosis before therapy; 7 [23%] developed fibrosis and 3 [10%] cirrhosis on treatment).
McHenry PM, Bingham EA, Callender ME, Delvin PB, O'Hara MD, Ferguson WR, Laird JD, et al. (1992). Dynamic hepatic scintigraphy in the screening of patients for methotrexate-induced hepatotoxicity. Br J Dermatol. (Among 63 patients with psoriasis having 87 dynamic scintigraphy scans during methotrexate therapy, 20 scans were abnormal, including 83% of 6 with moderate-severe fibrosis and 22% of 81 without fibrosis).
Weinblatt ME, Weissman BN, Holdsworth DE, Fraser PA, Maier AL, Falchuk KR, Coblyn JS. (1992). Long-term prospective study of methotrexate in the treatment of rheumatoid arthritis: 84-month update. Arthritis Rheum. (26 patients with rheumatoid arthritis enrolled in study of methotrexate [7.5-15 mg weekly], liver biopsies showed no fibrosis at 2 years [n=17; mean dose 1.1 g], one at 4 years [n=15; 2.0 g], and another at 6 years [n=10, 3.1 g]; both cases were Roenigk IIIA only, but both had normal biopsy previously).
Arias JM, Morton KA, Albro TE, Patch GG, Valdivia S, Greenberg HE, Christian PE, et al. (1993). Comparison of methods for identifying early methotrexate-induced hepatotoxicity in patients with rheumatoid arthritis. J Nucl Med. (Analysis of 16 patients undergoing 22 sets of noninvasive tests of liver disease while on methotrexate for 0.5 to 8 years; comparing 13 patients with minimal or no histologic changes to 9 patients with Roenigk II and III changes, liver enzymes were elevated in 0% vs 22%, aminopyrine breath tests 54% vs 55%, hepatic technetium scans 0% vs 11%; none being adequately sensitive and specific compared to liver biopsy).
Walker AM, Funch D, Dreyer NA, Tolman KG, Kremer JM, Alarcón GS, Lee RG, et al. (1993). Determinants of serious liver disease among patients receiving low-dose methotrexate for rheumatoid arthritis. Arthritis Rheum. (In a survey of 107 US rheumatologists, they identified 24 verifiable cases of cirrhosis attributable to methotrexate and compared them to 39 matched controls; patients with cirrhosis were older [54 vs 42 years], received a higher cumulative dose [1.9 vs 0.7 g], but did not differ by body weight, diabetes, sex, other medication use or recorded alcohol use; estimated rate of serious liver disease as 0.1% after 5 years of methotrexate use).
Minocha A, Dean HA, Pittsley RA. (1993). Liver cirrhosis in rheumatoid arthritis patients with long-term methotrexate. Vet Hum Toxicol. (Among 25 patients with rheumatoid arthritis undergoing 29 surveillance liver biopsies during methotrexate therapy [1-5 years], 1 had fibrosis and 2 cirrhosis [both had elevations in serum enzymes and were obese and diabetic]).
Brass EP. (1993). Hepatic toxicity of antirheumatic drugs. Cleve Clin J Med. (Short review of hepatotoxicity of nonsteroidals, salicylates, methotrexate, penicillamine and gold).
Nohlgård C, Rubio CA, Kock Y, Hammar H. (1993). Liver fibrosis quantified by image analysis in methotrexate-treated patients with psoriasis. J Am Acad Dermatol. (Sirius red staining on 46 liver biopsies from 26 patients with psoriasis analyzed by image analysis found higher percent of fibrosis in patients with psoriasis than controls [0.9%], but no correlation with methotrexate therapy, total dose, nor with Roenigk classification [Grade I with 11.4%, IIIA with 9.3%, IIIB 24% and IV 11.8%]).
Carvallo A, Wolff C, Armas R, Villanueva P, Donoso G, Náira N, Lobo G, et al. (1993). Rev Med Chil.
Lacki JK, Samborski W, Machiewicz SH. (1993). Transient increase of aminotransferases in RA patients treated with methotrexate. Z Rheumatol.
Shiroky JB, Neville C, Esdaile JM, Choquette D, Summer M, Hazeltine M, Bykerk V, et al. (1993). Low-dose methotrexate with leucovorin(folinic acid) in the management of rheumatoid arthritis. Results of a multicenter randomized, double-blind, placebo-controlled trial. Arthritis Rheum. (Among 92 patients with rheumatoid arthritis treated with methotrexate and either placebo or folinic acid, there were fewer side effects in those on folate [60% reduction in enzyme elevations] with no difference in efficacy).
McKendry RJ, Dale P. (1993). Adverse effects of low dose methotrexate therapy in rheumatoid arthritis. J Rheumatol. (Among 144 patients with rheumatoid arthritis starting methotrexate therapy, 75% stopped therapy before 5 years; 53% for adverse events, 14% for elevated liver tests, usually in first 2 years).
Morgan SL, Baggott JE, Vaughn WH, Austin JS, Veitch TA, Lee JY, Koopman WJ, et al. (1994). Supplementation with folic acid during methotrexate therapy for rheumatoid arthritis. A double-blind placebo-controlled trial. Ann Intern Med. (79 patients with rheumatoid arthritis treated with methotrexate were given placebo or 5 or 27.5 mg of folate weekly; efficacy was similar, but side effects were less with folate treatment, particularly at higher dose; also prevented folate deficiency which occurred by one year in placebo recipients).
Kremer JM Alarcon GS Lightfoot RW Wilkens RF Furst DE Willliams HJ Dent PB,
Kremer JM, Alarcón GS, Lightfoot RW, Willkens RF, Furst DE, Williams HJ, Dent PB, et al. (1994). Methotrexate for rheumatoid arthritis. Suggested guidelines for monitoring liver toxicity. Arthritis Rheum. (Review of hepatotoxicity of methotrexate in rheumatoid arthritis and delineation of guidelines; among 295 biopsies taken before therapy, only 3.7% had fibrosis and none cirrhosis, compared to fibrosis rates of 15% and cirrhosis of 0.3% on treatment; ALT elevations >2 times ULN occurred in 3.4% on methotrexate vs 0.4% on placebo or gold usually during first 2-3 years; recommend pretreatment biopsy only in patients with raised enzymes or risk factors for liver disease, regular liver test monitoring at 4-8 week intervals and repeat liver biopsy if AST elevations occur [at least 5] or albumin levels fall; discontinue if Roenigk grade IIIB or IV or if AST elevations present and unable to do liver biopsy).
Petrazzuoli M, Rothe MJ, Grin-Jorgensen C, Ramsey WH, Grant-Kels JM. (1994). Monitoring patients taking methotrexate for hepatotoxicity. J Am Acad Dermatol. (Survey of 70 gastroenterologists in practice; only 33% were monitoring patients with psoriasis or rheumatoid arthritis on methotrexate therapy).
Breithaupt H. (1994). Z Rheumatol.
Exadaktylos P, Reiss T, Schobess R, Hommann M, Höhne S, Beck A. (1994). Klin Padiatr.
Fabbri A, Motta E, Ferrari S, Longhi C, Marchi E, Bacci G, Figus E, et al. (1994). High-dose methotrexate treatment and liver function in patients with osteosarcoma. J Intern Med. (Among 14 patients with osteosarcoma who had received high dose methotrexate therapy [30-57 g/m^2^], galactose elimination decreased minimally while aminopyrine clearance and routine liver tests did not change between baseline and end of therapy).
Goodman TA, Polisson RP. (1994). Methotrexate: adverse reactions and major toxicities. Rheum Dis Clin North Am. (Review of side effects of methotrexate therapy in rheumatoid arthritis).
Schnabel A, Reinhold-Keller E, Willmann V, Gross WL. (1994). Tolerability of methotrexate starting with 15 or 25 mg/week for rheumatoid arthritis. Rheumatol Int. (Controlled trial of methotrexate starting at either 15 or 25 mg/week in 168 patients with rheumatoid arthritis found slightly higher side effects with higher initial dose, but similar withdrawal rates [~23%] at 12 months; ALT or AST elevations occurred in 38% starting with 15 mg/week and 44% with 25 mg/week).
Van Dooren-Greebe RJ, Kuijpers AL, Mulder J, De Boo T, Van de Kerkhof PC. (1994). Methotrexate revisited: effects of long-term treatment in psoriasis. Br J Dermatol. (Retrospective analysis of 113 patients with psoriasis treated with methotrexate [7.5-15 mg/week] for an average of 9 years [mean total dose 4.8 g]; methotrexate was discontinued in 71 patients, 12 [17%] for liver test abnormalities; 105 liver biopsies done in 55 patients, 7 [13%] had fibrosis and 2 [4%] cirrhosis with poor correlation with total dose, duration of therapy or abnormal liver tests).
Chandran G, Ahern MJ, Hall PD, Geddes R, Smith MD, Hill W, Harley JH. (1994). Cirrhosis in patients with rheumatoid arthritis receiving low dose methotrexate. Br J Rheumatol. (Three cases; 68-70 year old men with long standing rheumatoid arthritis treated with methotrexate for 5, 7 and 11 years [3.9, 7.2 and 10 g total dose] presented with varices or ascites; 2 had no alcohol use and all had minimally and only intermittently abnormal AST values during long term monitoring).
Bergquist SR, Felson DT, Prashker MJ, Freedberg KA. (1995). The cost-effectiveness of liver biopsy in rheumatoid arthritis patients treated with methotrexate. Arthritis Rheum. (Cost effectiveness of liver biopsy during methotrexate therapy was dependent on the likelihood of cirrhosis and was $52,000 per year of life saved at 10 years, but $1.9 million per year of life saved at 5 years).
Kremer JM, Kaye GI, Kaye NW, Ishak KG, Axiotis CA. (1995). Light and electron microscopic analysis of sequential liver biopsy samples from rheumatoid arthritis patients receiving long-term methotrexate therapy: follow up over long treatment intervals and correlation with clinical and laboratory variables. Arthritis Rheum. (Analysis of 170 liver biopsies from 27 patients with rheumatoid arthritis treated with methotrexate for 2 to 11 years [0.8-10.4 g]; there were minimal increases in average Roenigk score [1.8 at baseline to 2.3 at year 3 and 2.4 at year 6] and no significant change in semiquantitative estimates of electron microscopic features of fat, bile, collagen or smooth endoplasmic reticulum).
Oogarah PK, Rowland PL, Mitchell DM, Smith A, Chalmers RG, Rowan B, Haboubi NY. (1995). Abnormalities of serum type III procollagen aminoterminal peptide in methotrexate-treated psoriatic patients with normal liver histology do not correlate with hepatic ultrastructural changes. Br J Dermatol. (Electron microscopic analysis of liver biopsies described by Mitchell et al. [1990] showed no correlation of changes with PIIIP levels; collagen in space of Disse present in 82% of biopsies and amount did not correlate with light microscopic or PIIIP elevations).
al-Lamki Z, Thomas E, el-Banna N, Jaffe N. (1995). Acute urticaria and hepatitis complicating high-dose methotrexate therapy. Med Pediatr Oncol. (3.5 year old girl with osteosarcoma given 22 courses of methotrexate with leucovorin rescue with excellent response, but then had anaphylactic reaction with 23rd course with urticaria, facial edema, and jaundice [bilirubin 19.7 mg/dL, ALT 4278 U/L, LDH 10,968 U/L, protime 15.3 sec], resolving in 4 weeks with immediate erythema and nausea on brief methotrexate rechallenge).
Boffa MJ, Chalmer RJ, Haboubi NY, Shomaf M, Mitchell DM. (1995). Sequential liver biopsies during long-term methotrexate treatment for psoriasis: a reappraisal. Br J Dermatol. (Analysis of 124 liver biopsies taken from 49 patients with psoriasis treated with methotrexate; between the initial and last biopsy, 24% improved, 57% did not change and 18% worsened, but none developed cirrhosis and rates of fibrosis fell from 22% to 20% despite another average 2.4 g of methotrexate).
Erickson AR, Reddy V, Vogelgesang SA, West SG. (1995). Usefulness of the American College of Rheumatology recommendations for liver biopsy in methotrexate-treated rheumatoid arthritis. Arthritis Rheum. (Using the initial Psoriatic Task Force recommendations, 66 of 112 patients with rheumatoid arthritis treated with methotrexate underwent 110 liver biopsies and 5 were found to have advanced fibrosis or cirrhosis [Roenigk IIIB or IV], whereas applying the new American College of Rheumatology guidelines only 15 would have undergone 18 biopsies and 4 of the 5 with advanced fibrosis would have been identified, the case of cirrhosis missed being a patient with diabetes and perhaps deserving histological monitoring).
Lower EE, Baughman RP. (1995). Prolonged use of methotrexate for sarcoidosis. Arch Intern Med. (Among 50 patients with sarcoidosis treated with methotrexate for 2-6 years, liver biopsy histology became abnormal in 6 [15%], but findings were not reflected in serum enzyme elevations).
Reiff A, Shaham B, Wood BP, Bernstein BH, Stanley P, Szer IS. (1995). High dose methotrexate in the treatment of refractory juvenile rheumatoid arthritis. Clin Exp Rheumatol. (Use of higher doses of methotrexate in 21 children with severe juvenile rheumatoid arthritis was beneficial in only 33% of patients; transient ALT or AST elevations occurred in 38% and all resolved with holding dose, not requiring permanent discontinuation).
Tamaro G, Danek GM, Mangiarotti MA, Tamaro P, Zanazzo GA. (1995). Methotrexate therapy and liver fibrosis: are human prolyl hydroxylase and type IV collagen reliable and sensitive markers?. Int J Clin Lab Res. (Among 13 children with leukemia treated with high dose methotrexate, 62% had elevations in serum prolyl hydroxylase and type IV collagen, suggesting that these tests may identify patients with significant liver injury; but histological verification was not done).
Salaffi F, Carotti M, Sartini A, Cervini C. (1995). A prospective study of the long-term efficacy and toxicity of low-dose methotrexate in rheumatoid arthritis. Clin Exp Rheumatol. (Among 51 Italian patients with rheumatoid arthritis treated with methotrexate weekly for up to 3 years, 14% had transient ALT or AST elevations, all resolving spontaneously or with dose modification).
Franck H, Rau R, Herborn G. (1996). Thrombocytopenia in patients with rheumatoid arthritis on long-term treatment with low dose methotrexate. Clin Rheumatol. (Among 315 patients with rheumatoid arthritis treated with methotrexate, 13 developed thrombocytopenia [<100,000/μL], after 1-100 [mean=41] months of therapy [mean total dose 1.9 g], most instances improved when methotrexate or other medications were withdrawn).
ter Borg EJ, Seldenrijk CA, Timmer R. (1996). Liver cirrhosis due to methotrexate in a patient with rheumatoid arthritis. Neth J Med. (49 year old woman with rheumatoid arthritis underwent liver biopsy after ~8 years of methotrexate therapy [total dose 6 g] with ALT 52 U/L, Alk P 180 U/L, albumin 3.5 g/dL, and platelet count 76,000/μL; ultrasound showed splenomegaly; biopsy [previously normal] showing early cirrhosis; liver tests fell to normal on stopping methotrexate but platelets remained low [124,000/μL]).
Dufour JF, Kaplan MM. (1996). Methotrexate therapy and liver disease. N Engl J Med. (Patient with sclerosing cholangitis started on methotrexate had an increase in ALT [rising from 51 to 467 U/L] for two months, but a liver biopsy showed no change from earlier specimen and ALT levels subsequently fell to normal).
Furuya T, Totokawa S, Nakajima A, Suzuki T, Kashiwazaki S. (1996). Ryumachi.
Kawabe Y, Eguchi K, Tsuboi M, Kita M, Tsukada T, Takashima H, Mizokami A, et al. (1996). Ryumachi.
Malatjalian DA, Ross JB, Williams CN, Colwell SJ, Eastwood BJ. (1996). Methotrexate hepatotoxicity in psoriatics: report of 104 patients from Nova Scotia, with analysis of risks from obesity, diabetes and alcohol consumption during long term follow-up. Can J Gastroenterol. (Among 104 patients with psoriasis treated with methotrexate for 1-11 years undergoing 477 liver biopsies, 7% had mild fibrosis before treatment; 46% developed fibrosis [26% mild, 20% moderate] and 3% cirrhosis; progression to fibrosis correlating with diabetes, but not social alcohol intake).
Kugathasan S, Newman AJ, Dahms BB, Boyle JT. (1996). Liver biopsy findings in patients with juvenile rheumatoid arthritis receiving long-term, weekly methotrexate therapy. J Pediatr. (Nine children with juvenile rheumatoid arthritis treated for at least 3 years with weekly methotrexate [total dose 0.8-2.3 g] underwent liver biopsy and all were normal [Roenigk I], and only one had mild steatosis).
vanDooren-Greebe RJ, Kuijpers AL, Buijs WC, Kniest PH, Corstens FH, Nagengast FM, de Boo T, et al. (1996). The value of dynamic hepatic scintigraphy and serum aminoterminal propeptide of type III procollagen for early detection of methotrexate-induced hepatic damage in psoriasis patients. Br J Dermatol. (25 patients with psoriasis treated with methotrexate [total dose 0.2-11 g; mean 3.9 g] underwent liver biopsy, PIIIP testing and dynamic scintigraphy; only 1 patient had fibrosis [Roenigk IIIA] who had both an elevated PIIIP and abnormal scan).
Biasi D, Bambara LM, Carletto A, Casaril M, Capra F, Caramaschi P, Corrocher R. (1996). Effects on fibrogenesis markers of rheumatoid arthritis therapy with methotrexate. J Rheumatol. (Among 20 patients with rheumatoid arthritis treated with methotrexate for 1 year, PIIIP levels were slightly higher than controls before therapy but actually decreased on average during therapy, while laminin levels did not change).
Jaskiewicz K, Voigt H, Blakolmer K. (1996). Increased matrix proteins, collagen and transforming growth factor are early markers of hepatotoxicity in patients on long-term methotrexate therapy. J Toxicol Clin Toxicol. (76 liver biopsies from 36 patients with psoriasis treated with methotrexate for 1-5 years were studied by immunohistochemistry showing slight and progressive increases in laminin, fibronectin and collagen in biopsies, with minimal or no changes by light microscopy).
Rebora A. (1996). Is methotrexate liver toxicity modest worldwide?. Br J Dermatol. (Letter in response to Boffa et al. [1995] raising issue of hepatitis C contributing to apparent hepatotoxicity of methotrexate; reply by authors that HCV testing was not done but is rare in Manchester UK).
Weinblatt ME. (1996). Methotrexate in rheumatoid arthritis: toxicity issues. Br J Rheumatol. (Editorial on methotrexate hepatotoxicity and guidelines for monitoring).
Zachariae H, Sød H, Heickendorff L. (1996). Methotrexate-induced liver cirrhosis. Clinical, histological and serological studies - a further 10-year follow-up. Dermatology. (Long term follow up on 25 patients with psoriasis who developed cirrhosis on methotrexate therapy [reported in 1987]; the majority continued on lower doses of methotrexate and tolerated therapy well; 13 died, but only one of liver failure [all with autopsies had cirrhosis]; 13 appeared not to have cirrhosis on follow up liver biopsy and PIIIP levels were largely normal, suggesting that methotrexate induced cirrhosis is rarely progressive even with continuing therapy, at least at low doses).
Boffa MJ, Smith A, Chalmer RJG, Mitchell DM, Rowan B, Warnes TW, Shomaf M, et al. (1996). Serum type III procollagen aminopeptide for assessing liver damage in methotrexate-treated psoriasis patients. Br J Dermatol. (Serum PIIIP levels were measured at time of 147 liver biopsies in 87 patients with psoriasis on methotrexate; raised PIIIP levels found in 18% of 28 patients with a normal biopsy, 42% of 12 with steatosis, 54% of 26 with inflammation, 78% of 18 with fibrosis and 100% of 3 with cirrhosis; among 17 patients followed serially, elevations in PIIIP occurred in all 6 with progression vs only 3 of 11 without).
Kremer JM, Furst DE, Weinblatt ME, Blotner SD. (1996). Significant changes in serum AST across hepatic histological biopsy grades: prospective analysis of 3 cohorts receiving methotrexate therapy for rheumatoid arthritis. J Rheumatol. (Among 94 patients with rheumatoid arthritis treated with methotrexate who underwent 354 liver biopsies, AST levels were higher in those with higher Roenigk scores and elevations were associated with abnormal liver biopsy grade).
Bologna C, Viu P, Picot MC, Jorgensen C, Sany J. (1997). Long-term follow-up of 453 rheumatoid arthritis patients treated with methotrexate: an open retrospective, observational study. Br J Rheumatol. (Among 453 French patients with rheumatoid arthritis treated with methotrexate given weekly for an average of 3 years [0.3 to 9 years], 13% had elevated liver tests leading to withdrawal in 2.3%; no deaths from liver disease and no mention of cirrhosis or liver biopsies).
Beyeler C, Reichen J, Thomann SR, Lauterburg BH, Gerber NJ. (1997). Quantitative liver function in patients with rheumatoid arthritis treated with low-dose methotrexate: a longitudinal study. Br J Rheumatol. (Among 117 patients with rheumatoid arthritis treated with methotrexate and monitored yearly with galactose elimination, aminopyrine breath tests and bile acids, there was a decline in liver function tests with little correlation with routine test abnormalities; elevations in ALT occurred in 8%, GGT in 23%, bile acid levels in 2.4%; no correlation found between Roenigk score and decline in liver function tests in 16 patients with liver biopsy).
Hashkes PJ, Balistreri WF, Bove KE, Ballard ET, Passo MH. (1997). The long-term effect of methotrexate therapy on the liver in patients with juvenile rheumatoid arthritis. Arthritis Rheum. (Liver biopsies done on 14 children with juvenile rheumatoid arthritis treated with long term methotrexate found no fibrosis but minor changes found in 13, anisonucleosis, mild portal or lobular inflammation, and 3 with mild steatosis).
Kremer JM. (1997). Safety, efficacy, and mortality in a long-term cohort of patients with rheumatoid arthritis taking methotrexate: followup after a mean of 13.3 years. Arthritis Rheum. (Further follow up on initial cohort of 29 patients with rheumatoid arthritis [Kremer 1986] treated with long term methotrexate; 52% of patients remained on therapy for >10 years; 9 of the cohort had died, none of liver disease; among 10 still actively followed [mean total dose 9.7 g], none had clinically apparent liver disease).
Lewis JH. (1997). Monitoring for methotrexate hepatotoxicity in patients with rheumatoid arthritis: another hepatologist's perspective. J Rheumatol. (Editorial on methotrexate hepatotoxicity in rheumatoid arthritis endorsing the use of serial ALT and AST determinations to identify patients at risk of developing significant fibrosis during therapy and thus avoiding liver biopsy in most patients).
Stein CM, Brooks RH, Pincus T. (1997). Effect of combination therapy with cyclosporine and methotrexate on liver function test results in rheumatoid arthritis. Arthritis Rheum. (No differences in ALT elevations between patients on methotrexate alone [3%] vs its combination with cyclosporine [2%] for 24 weeks).
Kremer JM. (1997). Liver toxicity does not have to follow methotrexate therapy of patients with rheumatoid arthritis. Am J Gastroenterol. (Editorial on issue of monitoring patients with rheumatoid arthritis on methotrexate therapy suggested that frequent determinations of ALT and AST [at least 9 per year] allows for identification of patients at risk for developing progressive fibrosis; those with >50% of values elevated based upon results from Kremer et al. 1996).
West SG. (1997). Methotrexate hepatotoxicity. Rheum Dis Clin North Am. (Extensive review of methotrexate hepatotoxicity with discussion of both Psoriasis Task Force and American College of Rheumatology recommendations).
Ahern MJ, Smith MD, Roberts-Thomson PJ. (1998). Methotrexate hepatotoxicity: what is the evidence?. Inflamm Res. (Editorial on American College of Rheumatology recommendations for monitoring for liver injury during methotrexate therapy of rheumatoid arthritis, guidelines prudent but of unproven benefit).
Hakim NS, Kobienia B, Benedetti E, Bloomer J, Payne WD. (1998). Methotrexate-induced hepatic necrosis requiring liver transplantation in a patient with rheumatoid arthritis. Int Surg. (40 year old man with rheumatoid arthritis developed acute liver failure after 6 months of methotrexate therapy when he presented with rapid rise in ALT ["levels of several thousands"] and presence of HBsAg without anti-HBc in serum requiring liver transplantation, but no information on HBsAg status in follow up).
Narváez J, Rodriguez-Moreno J, Martinez-Aguilá MD, Clavaguera MT. (1998). Severe hepatitis linked to B virus infection after withdrawal of low dose methotrexate therapy. J Rheumatol. (67 year old man with rheumatoid arthritis treated with methotrexate [7.5 mg/week] and prednisone [5 mg/day] for 2 years [previous HBsAg status not known] developed acute hepatitis 3 weeks after stopping methotrexate because of pulmonary toxicity [bilirubin 1.8 mg/dL, ALT 252 U/L, Alk P 135 U/L, presence of HBsAg, IgM anti-HBc, anti-HBe, and HBV DNA], progressing to hepatic failure and death 6 months later).
Roenigk HH, Auerbach R, Maibach H, Weinstein G, Lebwohl M. (1998). Methotrexate in psoriasis: consensus conference. J Am Acad Dermatol. (Update of recommendations for use of methotrexate and monitoring for side effects; pretreatment liver biopsy recommended for patients with evidence of liver disease or significant risk factors; monitoring of liver chemistries every 4-8 weeks; liver biopsy on treatment after each 1.5 g of therapy and more frequent if liver tests are abnormal).
Burak KW, Urbanski SJ, Swain MG. (1998). Successful treatment of refractory type 1 autoimmune hepatitis with methotrexate. J Hepatol. (52 year old woman with refractory autoimmune hepatitis that worsened on azathioprine had a remission on methotrexate [7.5 mg/wk orally]).
Hashkes PJ, Balistreri WF, Bove KE, Ballard ET, Passo MH. (1999). The relationship of hepatotoxic risk factors and liver histology in methotrexate therapy for juvenile rheumatoid arthritis. J Pediatr. (Among 33 liver biopsies from 25 patients with juvenile rheumatoid arthritis treated with methotrexate for 1.5-12 years [total dose 0.5-8.4 g], 82% were normal and 6% had fibrosis [Roenigk IIIA only]; obesity and ALT or AST elevations were found to be risk factors for abnormal histology).
Locatelli M, Colleoni M, Noberasco C, Nolé F, Orlando L, Munzone E, Peruzzotti G, et al. (1999). Hepatic toxicity from cyclophosphamide, methotrexate, fluorouracil (CMF regimen). Ann Oncol. (Among 264 patients given methotrexate and fluorouracil intravenously twice monthly and oral cyclophosphamide for breast cancer, 40% had ALT elevations, 19% above 5 times ULN, but all resolved within 30 days).
Suzuki Y, Uehara R, Tajima C, Noguchi A, Ide M, Ichikawa Y, Mizushima Y, et al. (1999). Elevation of serum hepatic aminotransferases during treatment of rheumatoid arthritis with low-dose methotrexate. Risk factors and response to folic acid. Scand J Rheumatol. (Among 14 patients with rheumatoid arthritis treated with methotrexate who were started on folate [5 mg weekly, 36 hours after dosing], serum ALT levels fell in all within 3 months; two had exacerbations of arthritis and stopped folate).
Haustein UF, Rytter M. (2000). Methotrexate in psoriasis: 26 years' experience with low-dose long-term treatment. J Eur Acad Dermatol Venereol. (Retrospective analysis of clinical experience using methotrexate in 157 patients treated for up to 15 years [mean=5 years]; abnormal liver tests arose in 40 [25%] leading to stopping in 22 [14%], but no clinically apparent liver disease or cirrhosis).
Mok MY, Ng WL, Yuen MF, Wong RW, Lau CS. (2000). Safety of disease modifying anti-rheumatic agents in rheumatoid arthritis patients with chronic viral hepatitis. Clin Exp Rheumatol. (Among 29 Chinese patients with rheumatoid arthritis and chronic hepatitis [23 HBV; 6 HCV], ALT elevations occurred in 41% on hydroxychloroquine, 30% on methotrexate and 14% on gold vs 14% of 94 control patients without viral hepatitis).
Hirshberg B, Muszkat M, Schlesinger O, Rubinow A. (2000). Safety of low dose methotrexate in elderly patients with rheumatoid arthritis. Postgrad Med J. (Retrospective analysis of 33 patients with rheumatoid arthritis above age of 65 treated with methotrexate for at least 2 years; two patients stopped because of raised serum enzymes, but none developed clinically apparent liver injury).
Richard S, Guerret S, Gerard F, Tebib JG, Vignon E. (2000). Hepatic fibrosis in rheumatoid arthritis patients treated with methotrexate: application of a new semi-quantitative scoring system. Rheumatology. (Analysis of 74 liver biopsies from 57 patients with rheumatoid arthritis before or during methotrexate therapy using a new scoring system for fibrosis [graded at 4 sites giving scores of 0 to 35] found good correlation with Roenigk score, but no change in scores with methotrexate therapy).
Kuijpers AL, van de Kerkhof PC. (2000). Risk-benefit assessment of methotrexate in the treatment of severe psoriasis. Am J Clin Dermatol. (Review article on mechanism of action, pharmacology, efficacy and safety of methotrexate in psoriasis; in a study of 55 patients who underwent liver biopsy on therapy, 4% had cirrhosis and 13% fibrosis).
Lémann M, Zenjari T, Bouhnik Y, Cosnes J, Mesnard B, Rambaud J-C, Modigliani R, et al. (2000). Methotrexate in Crohn's disease: long-term efficacy and toxicity. Am J Gastroenterol. (Among 49 patients with Crohn disease treated with methotrexate for more than 6 months, serum enzyme elevations occurred in 10 leading to withdrawal in 2 patients; liver biopsies showed mild steatosis in 1 and mild fibrosis in two others).
Zachariae H. (2000). Liver biopsies and methotrexate: a time for reconsideration?. J Am Acad Dermatol. (Review of role of liver biopsy in monitoring methotrexate hepatotoxicity in patients with psoriasis and rheumatoid arthritis; PIIIP levels may provide a means of reducing number of biopsies, restricting surveillance biopsies to patients with high risk of having fibrosis).
Te HS, Schiano TD, Kuan SF, Hanauer SB, Conjeevaram HS, Baker AL. (2000). Hepatic effects of long-term methotrexate use in the treatment of inflammatory bowel disease. Am J Gastroenterol. (Among 32 patients with Crohn disease treated with methotrexate for 1-4 years, 20 underwent liver biopsy after 1.5-5.4 g of therapy given for 1-5 years; only 1 had fibrosis which was mild, and ALT and AST elevations were rare).
Weinblatt ME, Dixon JA, Falchuk KR. (2000). Serious liver disease in a patient receiving methotrexate and leflunomide. Arthritis Rheum. (51 year old man with rheumatoid arthritis was treated with leflunomide and methotrexate and had several ALT elevations and decline in platelet count during first 1-2 years of therapy and, after 3.5 years [total dose 4.5 g], a liver biopsy showed cirrhosis and mild steatosis without inflammation: Case 2).
Langman G, Hall PM, Todd G. (2001). Role of non-alcoholic steatohepatitis in methotrexate-induced liver injury. J Gastroenterol Hepatol. (Retrospective review of paired liver biopsies from 24 patients with methotrexate associated liver injury; 17 had features suggestive of nonalcoholic steatohepatitis [NASH] of whom 13 had risk factors such as obesity and diabetes).
Wollina U, Ständer K, Barta U. (2001). Toxicity of methotrexate treatment in psoriasis and psoriatic arthritis - short- and long-term toxicity in 104 patients. Clin Rheumatol. (Analysis of adverse events occurring in 104 patients with psoriasis treated with methotrexate for undefined period, ALT and AST elevations were the most frequent adverse event both during early and long term therapy).
van Ede AE, Laan RF, Rood MJ, Huizinga TW, van de Laar MA, van Denderene CJ, Westgeest TAA, et al. (2001). Effect of folic or folinic acid supplementation on the toxicity and efficacy of methotrexate in rheumatoid arthritis: a forty-eight week, multicenter, randomized, double-blind, placebo-controlled study. Arthritis Rheum. (Randomized controlled trial of folic acid [1 mg/day] vs folinic acid [7.5 mg/week] vs placebo in 434 patients with rheumatoid arthritis treated with methotrexate [7.5-25 mg/week] for 48 weeks, found higher toxicity related withdrawals with placebo [38%] compared to folate [17%] or folinic acid [12%]; elevated ALT levels occurred in 26% on placebo, 4% on folic acid and 4% on folinic acid; no differences in efficacy).
Venkataramani A, Jones MB, Sorrell MF. (2001). Methotrexate therapy for refractory chronic active autoimmune hepatitis. Am J Gastroenterol. (59 year old man with refractory autoimmune hepatitis and allergy to azathioprine had a biochemical remission on methotrexate [15 mg/wk]).
Zachariae H, Heickendorff L, Sogaard H. (2001). The value of amino-terminal propeptide of type III collagen in routine screening for methotrexate-induced liver fibrosis: a 10-year follow-up. Br J Dermatol. (Retrospective analysis of 70 patients with psoriasis on methotrexate therapy who were monitored with PIIIP levels after an initial liver biopsy; only 4 [6%] developed fibrosis, all of whom had elevations in PIIIP levels compared to only 2 of 66 who did not develop fibrosis).
Ito S, Nakazono K, Murasawa A, Mita Y, Hata K, Saito N, Kikuchi M, et al. (2001). Development of fulminant hepatitis B (precore variant mutant type) after the discontinuation of low-dose methotrexate therapy in a rheumatoid arthritis patient. Arthritis Rheum. (75 year old with rheumatoid arthritis and HBsAg carrier state [normal ALT and no HBeAg] was treated with methotrexate and prednisone for 3 years, but discontinued when ALT began to rise [112 U/L], and within a few weeks she presented with acute hepatitis [bilirubin 9.7 mg/dL, ALT 1016 U/L, prothrombin index 32%, presence of HBeAg and HBV DNA polymerase], dying of hepatic failure a few weeks later).
Cutolo M, Seriolo B, Pizzorni C, Craviotto C, Sulli A. (2002). Methotrexate in psoriatic arthritis. Clin Exp Rheumatol. (Review of status of methotrexate therapy in psoriatic arthritis, makes claim that folate therapy reduces efficacy of methotrexate).
Kumar B, Saraswat A, Kaur I. (2002). Short-term methotrexate therapy in psoriasis: a study of 197 patients. Int J Dermatol. (Retrospective review of 243 short term cycles of methotrexate therapy in 197 patients with psoriasis in India, with low rate of serum enzyme elevations [1.2%], and no evidence of progressive liver injury in 8 patients who underwent paired liver biopsy).
Lahdenne P, Rapola J, Ylijoki H, Haapasaari J. (2002). Hepatotoxicity in patients with juvenile idiopathic arthritis receiving longterm methotrexate therapy. J Rheumatol. (Among 10 patients with juvenile rheumatoid arthritis undergoing liver biopsy during methotrexate therapy, all had fat, 5 had inflammation but none had fibrosis; Roenigk scores were 1-2 only).
van Outryve S, Schrijvers D, van den Brande J, Wilmes P, Bogers J, van Marck E, Vermorken JH. (2002). Methotrexate-associated liver toxicity in a patient with breast cancer: case report and literature review. Neth J Med. (60 year old woman with breast cancer developed fatigue and mild ALT elevations [64 to 98 U/L] during cycles 2 to 4 of methotrexate-fluorouracil-cyclophosphamide, resolving when methotrexate was replaced by mitoxantrone; biopsy showed centrolobular fat and ballooning).
Choi HK, Hernan MA, Seeger JD, Robins JM, Wolfe F. (2002). Methotrexate and mortality in patients with rheumatoid arthritis: a prospective study. Lancet. (In a retrospective analysis of a large cohort of patients with rheumatoid arthritis, methotrexate use was associated with decrease in all-cause mortality and particularly cardiovascular).
Kwoh CK, Anderson LG, Greene JM, Johnson DA, O'Dell JR, Robbins ML, Roberts WN, et al., American College of Rheumatology Subcommittee on Rheumatoid Arthritis Guidelines. (2002). Guidelines for the management of rheumatoid arthritis: 2002 update. Arthritis Rheum. (Guidelines for management of rheumatoid arthritis; recommended serial monitoring during methotrexate therapy with routine liver tests and liver biopsy in those with risk factors of liver disease or persistent liver test abnormalities).
Ros S, Juanola X, Condom E, Cañas C, Riera J, Guardiola J, Del Blanco J, et al. (2002). Light and electron microscopic analysis of liver biopsy samples from rheumatoid arthritis patients receiving long-term methotrexate therapy. Scand J Rheumatol. (Analysis of liver biopsies by light and electron microscopy taken from 42 Spanish patients with rheumatoid arthritis before and after 4 years of methotrexate found mild fibrosis in 14% at baseline vs 12% at year 4; mild increase in steatosis, smooth endoplasmic reticulum, and number of lysosomes after therapy, but no change in amount of collagen in the space of Disse).
Penalva Polo JC, Gómez Andrés A, Vela P, Niveiro M. (2002). Rev Esp Enferm Dig.
Fathi NH, Mitros F, Hoffman J, Straniero N, Labreque D, Koehnke R, Furst DE. (2002). Longitudinal measurement of methotrexate liver concentrations does not correlate with liver damage, clinical efficacy, or toxicity during a 3.5 year double blind study in rheumatoid arthritis. J Rheumatol. (40 patients enrolled in a controlled trial of methotrexate in varying weekly oral doses underwent liver biopsy before and after 1, 2 and 3.5 years; at least one ALT abnormality occurred in ~50%, and AST ~25% of patients; the average Roenigk and "Iowa" histological scores did not change, but 13% developed some degree of fibrosis [none cirrhosis], abnormalities did not correlate with methotrexate concentrations in liver, use of folic acid, but some correlation was found between AST values and worsening of Iowa score).
Yazici Y, Erkan D, Paget SA. (2002). Monitoring methotrexate hepatic toxicity in rheumatoid arthritis: is it time to update the guidelines?. J Rheumatol. (Among 182 patients with rheumatoid arthritis treated with methotrexate, 17% had at least one abnormal liver test, but no instances of cirrhosis or clinically apparent liver disease arose; authors questioned the need of extensive monitoring).
Kremer JM. (2002). Not yet time to change the guidelines for monitoring methotrexate liver toxicity: they have served us well. J Rheumatol. (Review of the data that supported initial guidelines for monitoring serum enzymes during methotrexate therapy of rheumatoid arthritis suggesting that any elevation may be indicative of hepatic injury and that monitoring reduces occurrence of severe fibrosis).
Farrell GC. (2002). Drugs and steatohepatitis. Semin Liver Dis. (Hepatic changes similar to nonalcoholic steatohepatitis [NASH] occur with long term use of amiodarone, methotrexate and some nucleoside analogues; in contrast, corticosteroids, estrogens and tamoxifen appear to cause fatty liver by exacerbating pre-existing NASH).
Hoekstra M, van Ede AE, Haagsma CJ, van de Laar MAFJ, Huizinga TWJ, Kruijsen MWM, Laan RFJM. (2003). Factors associated with toxicity, final dose, and efficacy of methotrexate in patients with rheumatoid arthritis. Ann Rheum Dis. (Randomized trial of 48 weeks of methotrexate with or without folate supplementation in 411 patients with rheumatoid arthritis; ALT elevations >3 times ULN occurred in 26% of placebo vs 4% of folate supplemented groups; hepatotoxicity also more common with higher body weight index; folate did not affect efficacy but decreased withdrawals because of toxicity).
Hoekstra M, van de Laar MA, Bernelot Moens HJ, Kruijsen MW, Haagsma CJ. (2003). Longterm observational study of methotrexate use in a Dutch cohort of 1022 patients with rheumatoid arthritis. J Rheumatol. (Retrospective analysis of database on 1022 Dutch patients with rheumatoid arthritis treated with methotrexate, 64% remained on therapy for 5 and 50% after 9 years; factors favoring continuing therapy included folic acid supplementation; reason for stopping was liver test abnormalities in 14%).
Heydendael VMR, Spuls PhI, Opmeer BC, de Borgie CA, Saccozzi R, Luini A, Agullar M, et al. (2003). Methotrexate versus cyclosporine in moderate-to-severe chronic plaque psoriasis. N Engl J Med. (Controlled trial of 16 weeks of cyclosporine vs methotrexate in 88 patients with psoriasis found similar efficacy, but high dropout rate because of raised ALT levels in methotrexate group [27%]).
Vanhoof J, Landewe S, Van Wijngaerden E, Geusens P. (2003). High incidence of hepatotoxicity of isoniazid treatment for tuberculosis chemoprophylaxis in patients with rheumatoid arthritis treated with methotrexate or sulfasalazine and anti-tumour necrosis factor inhibitors. Ann Rheum Dis. (Among 88 patients with rheumatoid arthritis receiving disease modifying therapies, 8 were given isoniazid for latent tuberculosis half of whom developed hepatotoxicity, ALT levels rising to 82-330 U/L after 7-16 weeks and resolving 4-11 weeks after stopping; none were clinically apparent).
Baughman RP, Koehler A, Bejarano PA, Lower EE, Weber FL. (2003). Role of liver function tests in detecting methotrexate-induced liver damage in sarcoidosis. Arch Intern Med. (Among 68 patients with sarcoidosis undergoing 100 liver biopsies during 2-8 years of methotrexate therapy, 14% showed evidence of mild methotrexate toxicity, but no association found with ALT, AST or Alk P elevations or total dose).
Hytiroglou P, Tobias H, Saxena R, Abramidou M, Papadimitrian CS, Theise ND. (2004). The canals of Hering might represent a target of methotrexate hepatic toxicity. Am J Clin Pathol. (Analysis of 16 liver biopsies from 7 patients receiving methotrexate for psoriasis using special stains [cytokeratin 7] to identify the canals of Hering found a reduction of these structures in 13 patients with fibrosis due to methotrexate, the fibrosis following the distribution of the canals).
Boffa MJ. (2005). Methotrexate for psoriasis: current European practice. A postal survey. J Eur Acad Dermatol Venereol. (Survey of 69 European dermatologists on use of methotrexate in psoriasis; 59 [85%] used methotrexate but none requested baseline liver biopsies and <20% monitored patients with biopsies during therapy; among 10 fatalities attributed to methotrexate, 8 were caused by myelosuppression and two from liver failure).
Kent PD, Luthra HS, Michet C. (2004). Risk factors for methotrexate-induced abnormal laboratory monitoring results in patients with rheumatoid arthritis. J Rheumatol. (Retrospective chart review of 483 patients with rheumatoid arthritis treated with methotrexate [average 5 years], 4.6% of patients discontinued therapy because of liver test abnormalities, correlated with lack of folate supplementation, high BMI and untreated hyperlipidemia).
Whittle SL, Hughes RA. (2004). Folate supplementation and methotrexate treatment in rheumatoid arthritis: a review. Rheumatology. (Review of publications on folate supplementation during weekly methotrexate therapy of rheumatoid arthritis found no evidence that folate decreased efficacy, but clear evidence of fewer side effects including lower rates of ALT elevations; authors recommend 5 mg of folic acid weekly on the day after methotrexate is taken).
Kremer JM. (2004). Toward a better understanding of methotrexate. Arthritis Rheum. (Review of proposed mechanism of action and toxicity of methotrexate in autoimmune diseases; may cause increase in intracellular and extracellular adenosine levels which bind to its cellular membrane receptors and increase intracellular cyclic AMP which has immunosuppressive consequences).
Hagiyama H, Kubota T, Komano Y, Kurosaki M, Watanabe M, Miyasaka N. (2004). Fulminant hepatitis in an asymptomatic chronic carrier of hepatitis B virus mutant after withdrawal of low-dose methotrexate therapy for rheumatoid arthritis. Clin Exp Rheumatol. (72 year old with rheumatoid arthritis and HBsAg carrier state [normal ALT and no HBeAg] developed elevations in serum ALT [246 U/L] 2 years after starting methotrexate [4 mg/week] and prednisone [5 mg daily]; 2 months after stopping, she presented with acute liver failure [ALT 569 U/L, prothrombin index 65%, presence of HBeAg and HBV DNA] and died).
Ortiz-Alvarez O, Morishita K, Avery G, Green J, Petty RE, Tucker LB, Malleson PN, et al. (2004). Guidelines for blood test monitoring of methotrexate toxicity in juvenile idiopathic arthritis. J Rheumatol. (Monitoring liver enzymes in 89 children with juvenile rheumatoid arthritis at monthly intervals for an average of 3 years, identified 13 instances [15%] of ALT or AST elevations >2 times ULN, all resolved rapidly and methotrexate was either continued or restarted without recurrence).
Heydendael VM, Spuls PI, Bossuyt PM, Bos JD, de Rie MA. (2004). Analysis of risk factors in psoriatic patients with methotrexate-induced increases in transaminase levels. Arch Dermatol. (Reanalysis of high rate [28%] of ALT elevations in controlled trial of methotrexate vs cyclosporine A, inconclusive results).
Aithal GP, Haugk B, Das S, Card T, Burt AD, Record CO. (2004). Monitoring methotrexate-induced hepatic fibrosis in patients with psoriasis: are serial liver biopsies justified?. Aliment Pharmacol Ther. (Analysis of 121 biopsies from 66 patients with psoriasis treated with methotrexate for average of 5.4 years found advanced fibrosis arose in 2.6% of biopsies after 1.4-3 g, 8.2% after 4.5-6 g, and 32% after 10 g total dose; total number of cases uncertain; Roenigk score has less helpful than Ishak or Scheuer fibrosis scales).
Suissa S, Ernst P, Hudson M, Bitton A, Kezouh A. (2004). Newer disease-modifying antirheumatic drugs and the risk of serious hepatic adverse events in patients with rheumatoid arthritis. Am J Med. (Case control analysis of hepatic events in two US cohorts of 41,885 patients with rheumatoid arthritis treated with disease modifying agents, found no increase in cases of serious or non-serious events with leflunomide [rate ratio 0.9] compared to methotrexate, but higher rates with etanercept and infliximab [rate ratio 5.3]).
Gupta R, Gupta SK. (2005). Severe hepatotoxicity in a rheumatoid arthritis patient switched from leflunomide to methotrexate. MedGenMed. (44 year old woman with rheumatoid arthritis found to have elevated ALT [341 U/L] 9 months after starting leflunomide, resolving within 2 months of stopping, but recurring after 3 months of oral methotrexate which was tolerated for many years in the past [bilirubin 3.5 mg/dL, ALT 1297 U/L], resolving within 4 weeks of stopping).
Kinder AJ, Hassell AB, Brand J, Brownfield A, Grove M, Shadforth MF. (2005). The treatment of inflammatory arthritis with methotrexate in clinical practice: treatment duration and incidence of adverse drug reactions. Rheumatology (Oxford). (Among 673 patients with rheumatic diseases treated with methotrexate between 1986 and 1999, 74% continued on therapy for 5 years or more; 37 patients stopped because of abnormal liver tests; 25 patients died, but none from liver disease).
Mathew J, Leong MY, Morley N, Burt AD. (2005). A liver fibrosis cocktail? Psoriasis, methotrexate and genetic hemochromatosis. BMC Dermatol. (Two patients with hemochromatosis and psoriasis on long term methotrexate had minor abnormalities on liver biopsy without fibrosis).
Nieminen U, Höök-Nikanne J, Kärkäinen P, Niemelä S. (2005). Duodecim.
Yazici Y, Erkan D, Harrison MJ, Nikolov NP, Paget SA. (2005). Methotrexate use in rheumatoid arthritis is associated with few clinically significant liver function test abnormalities. Clin Exp Rheumatol. (Retrospective analysis of 182 patients with rheumatoid arthritis treated with methotrexate between 1985-1999; 16.5% had at least 1 abnormal ALT or AST, but only 2 discontinued drug for these findings and no patient developed clinically apparent liver injury; routine liver biopsies were not done).
Yazici Y, Sokka T, Kautiainen H, Swearingen C, Kulman I, Pincus T. (2005). Long term safety of methotrexate in routine clinical care: discontinuation is unusual and rarely the result of laboratory abnormalities. Ann Rheum Dis. (Among 248 patients with rheumatoid arthritis treated with methotrexate, 79% continued for at least 5 years; AST elevations occurred in 7% per year, but usually transient and <2 times ULN, none requiring permanent discontinuation).
Zachariae H. (2005). Have methotrexate-induced liver fibrosis and cirrhosis become rare? A matter for reappraisal of routine liver biopsies. Dermatology. (Editorial on issue of monitoring for liver fibrosis in patients with psoriasis on methotrexate; rates of cirrhosis in treated patients have decreased but major rates of cirrhosis were in those treated for >10 years, often with other hepatotoxic exposures).
Thomas JA, Aithal GP. (2005). Monitoring liver function during methotrexate therapy for psoriasis. Are routine biopsies really necessary?. Am J Clin Dermatol. (Review of role liver biopsy in monitoring patients with psoriasis on low dose methotrexate therapy; authors recommend pretreatment liver biopsy only in patients with evidence for liver disease or risk factors and routine surveillance biopsy only after total dose of 4 g, and use of Ishak or Scheuer fibrosis staging systems rather than Roenigk scale).
Maurice PD, Maddox AJ, Green CA, Tatnall F, Schofield JK, Stott DJ. (2005). Monitoring patients on methotrexate : hepatic fibrosis not seen in patients with normal serum assays of aminoterminal peptide of type III procollagen. Br J Dermatol. (Among 38 patients with psoriasis on methotrexate undergoing 70 liver biopsies and routine PIIIP testing, 4 patients had fibrosis and all 4 had at least one abnormal PIIIP level as did half of patients with normal liver biopsies; in 23 patients undergoing 2 biopsies, 4 worsened and all 4 had at least one abnormal PIIIP as did 63% of patients with no change; 46% of patients had persistently normal PIIIP values and none had fibrosis or worsening histology and might have avoided need for liver biopsy).
Chalmers RJG, Kirby B, Smith A, Burrows P, Little R, Horan M, Hextall JM, et al. (2005). Replacement of routine liver biopsy by procollagen III aminopeptide for monitoring patients with psoriasis receiving long-term methotrexate: a multicentre audit and health economic analysis. Br J Dermatol. (Comparison of costs between UK centers using PIIIP monitoring versus routine liver biopsy at different total methotrexate doses suggested seven-fold decrease in need for liver biopsy with serum fibrosis marker).
Berends MA, Snoek J, de Jong EM, van de Kerkhof PC, van Oijen MG, van Krieken JH, Drenth JP. (2006). Liver injury in long-term methotrexate treatment in psoriasis is relatively infrequent. Aliment Pharmacol Ther. (125 patients with psoriasis treated with methotrexate for average of 4.4 years underwent 278 liver biopsies; 71% did not change from baseline; 15% developed fibrosis including 2% with cirrhosis; poor correlation of fibrosis with ALT and AST elevations; over half had risk factors such as obesity, diabetes or alcohol use).
Khan S, Subedi D, Chowdhury MMU. (2006). Use of amino terminal type III procollagen peptide(P3MP) assay in methotrexate therapy for psoriasis. Postgrad Med J. (Retrospective analysis on 15 patients with psoriasis on long-term methotrexate who had abnormal PIIIP levels and underwent liver biopsy; one showing cirrhosis and two fibrosis).
Goujon C, Bérd F, Dahel K, Guillot I, Hennino A, Nosbaum A, Saad N, et al. (2006). Methotrexate for the treatment of adult atopic dermatitis. Eur J Dermatol. (20 patients with atopic dermatitis were treated with methotrexate, 15 having a response at 3 months and continuing therapy [7.5-25 mg/week], 10% had serum enzyme elevations, but none required stopping).
La Montagna G, Tirri R, Vitello R, Malesci D, Buono R, Mennillo G, Valentini G. (2006). Reumatismo. (Among 224 patients with rheumatoid arthritis treated with methotrexate for an average of 4 years, 9 [4%] had ALT or AST elevations requiring discontinuation).
Tilling L, Townsend S, David J. (2006). Methotrexate and hepatic toxicity in rheumatoid arthritis and psoriatic arthritis. Clin Drug Investig. (Prospective study of 550 patients with rheumatoid arthritis and 69 with psoriasis treated with methotrexate [1-30 mg/week] for up to 13 years [mean=3 years], rise in ALT or AST to >3 times ULN occurred in 14.5% of psoriasis vs 7.5% of rheumatoid arthritis patients; differences and most abnormalities were not explained by differences in alcohol use).
Berends MA, van Oijen MG, Snoek J, van de Kerkhof PC, Drenth JP, Han van Krieken J, de Jong EM. (2007). Reliability of the Roenigk classification of liver damage after methotrexate treatment for psoriasis: a clinicopathologic study of 160 liver biopsy specimens. Arch Dermatol. (Among 160 liver biopsies from 95 patients with psoriasis treated with oral methotrexate, reading for Roenigk score gave highly concordant results with initial local readings).
Correa G H, Paredes S N. (2007). Rev Med Chil. (Among 63 patients with psoriasis treated with methotrexate in Chile, 32% had elevation in liver tests; 10% had ALT values above 2 times ULN [97-321 U/L], most were transient, one resolved rapidly with stopping).
Gwak GY, Koh KC, Kim HY. (2007). Fatal hepatic failure associated with hepatitis B virus reactivation in a hepatitis B surface antigen-negative patient with rheumatoid arthritis receiving low dose methotrexate. Clin Exp Rheumatol. (59 year old woman with rheumatoid arthritis [with anti-HBs without HBsAg] who was treated with methotrexate [10 mg/week] and prednisone [5 mg/day] for 7 years developed acute hepatitis B reactivation [bilirubin 5.7 rising to 29.5 mg/dL, ALT 378 U/L, INR 3.4, presence of HBsAg, HBeAg and HBV DNA ~15 million copies/mL], progressing to hepatic failure and death within 8 weeks of onset).
Shimada K, Matsui T, Kawakami M, Nakayama H, Ozawa Y, Mitomi H, Tohma S. (2007). Methotrexate-related lymphomatoid granulomatosis: a case report of spontaneous regression of large tumours in multiple organs after cessation of methotrexate therapy in rheumatoid arthritis. Scand J Rheumatol. (54 year old woman with rheumatoid arthritis on methotrexate for 10 years presented with widespread lymphomatoid granulomatosis which spontaneously disappeared 3 months after stopping methotrexate).
Ting TV, Hashkes PJ. (2007). Methotrexate/naproxen-associated severe hepatitis in a child with juvenile idiopathic arthritis. Clin Exp Rheumatol. (2 year old girl with idiopathic arthritis treated with methotrexate and naproxen for 8 months had elevated AST [88 rising to 2372 U/L] with lethargy, hypoglycemia and high ammonia but normal bilirubin and INR and rapid recovery upon stopping methotrexate).
Saag KG, Teng GG, Patkar NM, Anuntiyo J, Finney C, Curtis JR, Paulus HE, et al., American College of Rheumatology. (2008). American College of Rheumatology 2008 recommendations for the use of nonbiologic and biologic disease-modifying antirheumatic drugs in rheumatoid arthritis. Arthritis Rheum. (Recommendations on use of disease modifying agents in rheumatoid arthritis including monitoring for liver disease).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no case was attributed to methotrexate).
Carneiro SC, Cássia FF, Lamy F, Chagas VL, Ramos-e-Silva M. (2008). Methotrexate and liver function: a study of 13 psoriasis cases treated with different cumulative dosages. J Eur Acad Dermatol Venereol. (13 Brazilian patients with psoriasis underwent liver biopsy before and after 1-4 g of oral methotrexate therapy; fibrosis found in none of 18 who received <2 g, in 1 of 7 after 3 g, and 2 of 4 after 4 g including 2 with cirrhosis; no mention of folate supplementation).
Cheng KK. (2008). Association of plasma methotrexate, neutropenia, hepatic dysfunction, nausea/vomiting and oral mucositis in children with cancer. Eur J Cancer Care(Engl). (Case control study in 28 children with leukemia given high dose iv methotrexate [5-12 g/m^2^]; found those with mucositis had higher serum methotrexate levels, but similar rates of ALT or AST elevations as those without mucositis).
Domènech E, Mañosa M, Navarro M, Masnou H, Garcia-Planella E, Zabana Y, Cabré E, et al. (2008). Long-term methotrexate for Crohn's disease: safety and efficacy in clinical practice. J Clin Gastroenterol. (Retrospective analysis of 44 patients with Crohn disease treated with methotrexate for average of 2 years [total dose 1.2 g]; ALT or AST elevations developed in 30% of patients requiring stopping therapy in 7%, but none developed cirrhosis or clinically apparent liver injury).
Hartmann U, Schmitt S, Reuss-Borst M. (2008). Z Rheumatol. (Case report of apparent autoimmune hepatitis arising in 17 year old woman with rheumatoid arthritis after 18 months of leflunomide therapy, controlled with prednisone and azathioprine).
Laharie D, Terrebonne E, Vergniol J, Chanteloup E, Chabrun E, Couzigou P, de Ledinghen V. (2008). Gastroenterol Clin Biol. (Review of hepatotoxicity of methotrexate).
Lapalus MG, Hot A, Fontana A, Guillaud O, Miossec P, Xcozaec J-Y, Dumorteir J. (2008). Epstein Barr virus-induced hepatitis associated with methotrexate treatment. J Clin Gastroenterol. (62 year old woman with systemic lupus on methotrexate and prednisone developed ascites [bilirubin 0.5 mg/dL, ALT 42 U/L, Alk P 85 U/L, albumin 3.1 and IgM anti-EBV], biopsy showing cirrhosis and "superimposed acute hepatitis", ultimately resolving).
Prey S, Paul C. (2009). Effect of folic or folinic acid supplementation on methotrexate-associated safety and efficacy in inflammatory disease: a systematic review. Br J Dermatol. (Systematic review of 6 studies of folic or folinic acid supplementation [648 patients] during methotrexate therapy of rheumatoid arthritis [n=5] or psoriasis [n=1]; significant reduction in liver adverse events by 36%, but not on other side effects and no difference between folinic or folic acid; whether folate supplemental affects effectiveness of methotrexate could not be assessed adequately).
Taylor WJ, Korendowych E, Nash P, Helliwell PS, Choy E, Krueger GG, Soriano ER, et al. (2008). Drug use and toxicity in psoriatic disease: focus on methotrexate. J Rheumatol. (Survey of rheumatologists regarding use of methotrexate in psoriasis and rheumatoid arthritis found a wide variability in practice of monitoring; use of folate was not assessed; 40 respondents had observed a case of cirrhosis due to methotrexate).
Dwyer N, Jones G, Kilpatrick D. (2009). Severe hepatotoxicity in a patient on bosentan upon addition of methotrexate: reversible with resumption of methotrexate without bosentan. J Clin Rheumatol. (45 year old with scleroderma on bosentan therapy developed liver test abnormalities 4 months after starting escalating doses of methotrexate [bilirubin 9.5 mg/dL, ALT 1189 U/L, Alk P 550 U/L, INR 1.3], resolving in 1 month of stopping both drugs; later tolerated methotrexate alone).
Katchamart W, Trudeau J, Phumethum V, Bombardier C. (2009). Efficacy and toxicity of methotrexate (MTX) monotherapy versus MTX combination therapy with non-biological disease-modifying antirheumatic drugs in rheumatoid arthritis: a systematic review and meta-analysis. Ann Rheum Dis. (Systematic review of 19 trials comparing methotrexate alone to its combination with other disease modifying agents in 2025 patients showed no improvement in efficacy by addition of other agents to methotrexate, but an increase in toxicity with combination therapy, including increased frequency of ALT elevations).
Lindsay K, Fraser AD, Layton A, Goodfield M, Gruss H, Gough A. (2009). Liver fibrosis in patients with psoriasis and psoriatic arthritis on long-term, high cumulative dose methotrexate therapy. Rheumatology (Oxford). (Retrospective analysis of liver biopsies in 54 patients with psoriasis treated with methotrexate for an average of 7 years; mild fibrosis [IIIA] was found in 22% of patients, but none had cirrhosis; history of alcohol use and PIIIP levels did not predict presence of fibrosis).
Boffa MJ, Smith A, Chalmers RJ. (2009). Comment on: Liver fibrosis in patients with psoriasis and psoriatic arthritis on long-term, high cumulative dose methotrexate therapy. Rheumatology (Oxford). (Letter in response to Lindsay et al. [2009] suggesting that serial normal PIIIP values in patients with psoriasis on methotrexate are helpful in providing reassurance that ongoing liver fibrosis will not be missed; response by authors suggests that more studies are needed).
Lu LJ, Bao CD, Dai M, Teng JL, Fan W, Du F, Yang NP, et al. (2009). Multicenter, randomized, double-blind, controlled trial of treatment of active rheumatoid arthritis with T-614 compared with methotrexate. Arthritis Rheum. (T-614, a novel immunomodulatory agent, was compared to methotrexate in a randomized controlled trial of 24 weeks in 489 patients with rheumatoid arthritis; similar efficacy; ALT elevations occurred in 24% on methotrexate vs 6% to 13.5% on T-614).
Neves C, Jorge R, Barcelos A. (2009). Acta Rheumatol Port. (Systematic review of methotrexate toxicities).
Periáñez-Párraga L, Pérez-Rodríguez O, do Pazo-Oubiña F, Crespí-Monjo M. (2009). Farm Hosp. (12 year old boy with acute leukemia developed raised ALT and bilirubin during high dose methotrexate therapy attributed to concurrent renal toxicity, resolving rapidly).
Salliot C, van der Heijde D. (2009). Long-term safety of methotrexate monotherapy in patients with rheumatoid arthritis: a systematic literature research. Ann Rheum Dis. (Systematic review of 21 prospective studies [3463 patients] on the safety of methotrexate in rheumatoid arthritis; using average dose of 9 mg/week for 3 years, 73% had at least one adverse event and 18.5% had a liver related event; overall in 769 patients followed prospectively, 20% had at least one elevation in liver enzymes, 13% above 2 times ULN, and 3.7% discontinued therapy for this reason).
Varatharajan N, Lim IG, Anandacoomarasamy A, Russo R, Byth K, Spencer DG, Manolios N, et al. (2009). Methotrexate: long-term safety and efficacy in an Australian consultant rheumatology practice. Intern Med J. (Retrospective analysis of outcomes of methotrexate therapy in 790 patients with chronic arthritis; therapy stopped in 18 patients [2%] because of liver test abnormalities, but no one developed cirrhosis or died of liver disease).
Ongaro A, De Mattei M, Della Porta MG, Rigolin G, Ambrosio C, Di Raimondo F, Pellati A, et al. (2009). Gene polymorphisms in folate metabolizing enzymes in adult acute lymphoblastic leukemia: effects on methotrexate-related toxicity and survival. Haematologica. (Polymorphisms of the two genes involved in folate metabolism correlated with an increased rate of hepatotoxicity [odds ratio 4.6 and 5.2] which was 29% overall; no correction was made for the multiple comparisons).
Amital H, Arnson Y, Chodick G, Shalev V. (2009). Hepatotoxicity rates do not differ in patients with rheumatoid arthritis and psoriasis treated with methotrexate. Rheumatology (Oxford). (Retrospective analysis of a health management organization records on 119 patients with rheumatoid arthritis and 690 with psoriasis treated with methotrexate showing that 45% of patients had at least one abnormal liver test, with no difference in rates of AST elevation between the two diagnostic groups).
Collin B, Vani A, Ogboli M, Moss C. (2009). Methotrexate treatment in 13 children with severe plaque psoriasis. Clin Exp Dermatol. (Retrospective analysis of 13 children with severe psoriasis treated with methotrexate for 6 weeks to 5 years [total dose 0.04-3.6 g]; 9 had transient and mild ALT elevations and 1 discontinued therapy after 6 weeks when ALT rose to 516 U/L).
Lynch M, Kirby B. (2010). Comment on: Hepatotoxicity rates do not differ in patients with rheumatoid arthritis and psoriasis treated with methotrexate. Rheumatology(Oxford). (Another letter in response to Amital [2009] arguing that standard liver tests alone are insufficient in monitoring for potential hepatotoxicity).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, methotrexate accounted for 134 cases [ranking 5th] with an adjusted risk odds ratio of 4.2).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, none of which were thought to be due to methotrexate).
Curtis JR, Beukelman T, Onofrei A, Cassell S, Greenberg JD, Kavanaugh A, Reed G, et al. (2010). Elevated liver enzyme tests among patients with rheumatoid arthritis or psoriatic arthritis treated with methotrexate and/or leflunomide. Ann Rheum Dis. (In a large, observational US database, ALT or AST elevations found in 17% of patients on leflunomide alone, 22% on methotrexate alone, and 31% on both; levels >2 times ULN in only 2% vs 1% vs 5% [on both]; risk factors for elevations were methotrexate dose, history of liver disease and alcohol use [1-2 drinks/day]).
Toscano E, Cotta J, Robles M, Lucena MA, Andrade RJ. (2010). Gastroenterol Hepatol. (Review of hepatotoxicity of different immunosuppressive agents including methotrexate).
Fournier MR, Klein J, Minuk GY, Bernstein CN. (2010). Changes in liver biochemistry during methotrexate use for inflammatory bowel disease. Am J Gastroenterol. (Among 87 patients with inflammatory bowel disease treated with methotrexate for an average of 2 years, 24% had liver test abnormalities, but most resolved without dose modification and no fibrosis or cirrhosis were found in liver biopsies from 20 patients).
Rogler G. (2010). Gastrointestinal and liver adverse effects of drugs used for treating IBD. Best Pract Res Clin Gastroenterol. (Review of recent literature on adverse effects of drugs used to treat inflammatory bowel disease including sulfasalazine, thiopurines, methotrexate, cyclosporine and tacrolimus).
Triantafyllou K, Vlachogiannakos J, Ladas SD. (2010). Gastrointestinal and liver side effects of drugs in elderly patients. Best Pract Res Clin Gastroenterol. (Review of drug adverse events in the elderly; injury seems to be more severe in older subjects, but frequency has not been proven to be increased and elderly may be at increased risk of hepatic fibrosis caused by methotrexate perhaps due to impaired renal function and frequent use of other medications).
Attar SM. (2010). Adverse effects of low dose methotrexate in rheumatoid arthritis patients. A hospital-based study. Saudi Med J. (Abstract: Among 71 patients with rheumatoid arthritis treated with methotrexate, 14% developed liver tests elevations).
Khokhar OS, Lewis JH. (2010). Hepatotoxicity of agents used in the management of inflammatory bowel disease. Dig Dis. (Review of hepatotoxicity of drugs used to treat inflammatory bowel disease including sulfasalazine, thiopurines, methotrexate and anti-TNF agents).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, 1% were hepatic and most common agents were isotretinoin, acetaminophen, valproic acid, carbamazepine, methotrexate, minocycline, lamotrigine, zidovudine, pemoline and ceftriaxone).
Barker J, Horn E, Lebwohl M, Warren R, Nast A, Rosenberg W, Smith C, International Psoriasis Council. (2011). Assessment and management of methotrexate hepatotoxicity in psoriasis patients: report from a consensus conference to evaluate current practice and identify key questions toward optimizing methotrexate use in the clinic. J Eur Acad Dermatol Venereol. (Review of the issue of hepatotoxicity of methotrexate and the reliability of monitoring with comparison of US, UK, European Union, German and Dutch guidelines; folate supplementation is recommended by most; pattern of details of monitoring and use of liver biopsy is variable and there is clearly a need for more accurate and less invasive means of assessing liver injury during methotrexate therapy).
Scientific Registry of Transplant Recipients. January 31, 2010. (Among 46,633 liver transplants done in the US between 2000 and 2009 in the SRTR registry, 31 [<0.1%] had the primary diagnosis of methotrexate induced cirrhosis).
Aithal GP. (2011). Medscape. Hepatotoxicity related to antirheumatic drugs. Nat Rev Rheumatol. (Review of hepatotoxicity of drugs used in rheumatic diseases; methotrexate causes ALT elevations and fibrosis in variable proportions of patients, more common in those with alcohol use, obesity, hyperlipidemia, metabolic syndrome and NASH).
Sultan MI, Biank VF, Telega GW. (2011). Successful treatment of autoimmune hepatitis with methotrexate. J Pediatr Gastroenterol Nutr. (Two girls, ages 7 and 11 years with autoimmune hepatitis refractory to therapy were switched from azathioprine to methotrexate [10 mg/wk subcutaneously] and had a complete biochemical response allowing eventual discontinuation of prednisone and maintained remission for more than 5 years on methotrexate alone).
Barbero-Villares A, Mendoza J, Trapero-Marugan M, Gonzalez-Alvaro I, Daudén E, Gisbert JP, Moreno-Otero R. (2011). Evaluation of liver fibrosis by transient elastography in methotrexate treated patients. Med Clin (Barc). (Among 53 patients with autoimmune diseases being treated with methotrexate [for 2 weeks to 10 years], transient elastography was abnormal in 4 [8%], but did not correlate with duration of therapy or total dose; liver histology was not studied).
Montaudié H, Sbidian E, Paul C, Maza A, Gallini A, Aractingi S, Aubin F, et al. (2011). Methotrexate in psoriasis: a systematic review of treatment modalities, incidence, risk factors and monitoring of liver toxicity. J Eur Acad Dermatol Venereol. (Systematic review of literature on hepatotoxicity of methotrexate in psoriasis identified 23 studies; "published studies do not confirm the incidence of hepatic fibrosis", the rate varying from 6-71% in 5 studies of 22-96 patients each followed for 1-11 years).
Moreno-Otero R, García-Buey L, García-Sanchez A, Trapero-Marugán M. (2011). Autoimmune hepatitis after long-term methotrexate therapy for rheumatoid arthritis. Curr Drug Saf. (57 year old man with rheumatoid arthritis developed jaundice 3 years after starting long term methotrexate [bilirubin 3.3 mg/dL, ALT 1715 U/L, Alk P 167 U/L, ANA 1:160 and previously negative], responding to corticosteroid therapy which was later stopped without relapse; unclear whether methotrexate was stopped).
Bishnoi P, Kumari R, Thappa DM. (2011). Monitoring methotrexate hepatotoxicity in psoriasis. Indian J Dermatol Venereol Leprol. (Review of safety and efficacy of methotrexate in psoriasis).
Gupta R, Bhatia J, Gupta SK. (2011). Risk of hepatotoxicity with add-on leflunomide in rheumatoid arthritis patients. Arzneimittelforschung. (Among 46 patients with rheumatoid arthritis who had leflunomide added to conventional disease modifying therapies, 22% had ALT or AST elevations, but none developed clinically apparent liver injury).
Anelli MG, Scioscia C, Grattagliano I, Lapadula G. (2012). Old and new antirheumatic drugs and the risk of hepatotoxicity. Ther Drug Monit. (Review of currently used antirheumatic drugs and their potential for hepatotoxicity).
Santiago García D, Saturansky E, Poncino D, Ortiz V, Martínez Artola Y, Rosenberg S, Abritta G, Palermo C, Enriquez N, Cravero A. (2012). Acta Gastroenterol Latinoam. (Among 118 patients with inflammatory arthritis, 47 [40%] had evidence of liver disease, including 35 [30%] with nonalcoholic fatty liver and 15 [13%] drug induced liver injury).
Tugnet N, Cooper SC, Douglas KM. (2012). Methotrexate therapy, rheumatoid arthritis, and life-threatening liver complications: should we be monitoring more closely?. Scand J Rheumatol. (26 year old woman with rheumatoid arthritis developed variceal hemorrhage after 4 years of methotrexate therapy [bilirubin 4.1 mg/dL, ALT 377 U/L, Alk P 166 U/L, platelets 80,000/μL, INR 2.4], improving after stopping and switching to etanercept).
Gilani ST, Khan DA, Khan FA, Ahmed M. (2012). Adverse effects of low dose methotrexate in rheumatoid arthritis patients. J Coll Physicians Surg Pak. (Methotrexate levels and clinical toxicity in 140 patients with rheumatoid arthritis on 10 mg/week found ALT or AST elevations in 2.1% and higher toxicity in those with higher levels in plasma).
Khan N, Abbas AM, Whang N, Balart LA, Bazzano LA, Kelly TN. (2012). Incidence of liver toxicity in inflammatory bowel disease patients treated with methotrexate: a meta-analysis of clinical trials. Inflamm Bowel Dis. (Metaanalysis of trials of methotrexate for inflammatory bowel disease identified 13 trials with 632 participants treated for 2.7-18 months; risk of ALT elevations [>2 times ULN] was 0.9 per 100 person-months).
Dávila-Fajardo CL, Swen JJ, Cabeza Barrera J, Guchelaar HJ. (2013). Genetic risk factors for drug-induced liver injury in rheumatoid arthritis patients using low-dose methotrexate. Pharmacogenomics. (Review of pharmacogenomics of methotrexate toxicity focusing upon MTHFR).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, one of which was attributed to methotrexate).
van Swelm RP, Laarakkers CM, Kooijmans-Otero M, de Jong EM, Masereeuw R, Russel FG. (2013). Biomarkers for methotrexate-induced liver injury: urinary protein profiling of psoriasis patients. Toxicol Lett. (Analysis of urinary protein profiles of patients on long term methotrexate therapy for psoriasis identified several urinary proteins that might serve as noninvasive markers of fibrosis progression including N-cadherin, ITIH4, haptoglobin and serotransferrin).
Ng LC, Lee YY, Lee CK, Wong SM. (2013). A retrospective review of methotrexate-induced hepatotoxicity among patients with psoriasis in a tertiary dermatology center in Malaysia. Int J Dermatol. (Among 66 patients with psoriasis treated with methotrexate between 2000 and 2009 at a Malaysian medical center, 58% had ALT or AST elevations during treatment, but therapy was stopped for enzyme elevations in only 6 patients and no patient developed cirrhosis).
Dávila-Fajardo CL, Swen JJ, Cabeza Barrera J, Guchelaar HJ. (2013). Genetic risk factors for drug-induced liver injury in rheumatoid arthritis patients using low-dose methotrexate. Pharmacogenomics. (Review of literature on clinical and genetic risk factors for methotrexate hepatotoxicity, mentions routine factors of obesity, alcohol use, diabetes, lack of folate supplementation, concurrent hepatotoxic medications, duration of therapy and total dose, and polymorphisms of the MTHFR gene, the role of which is not well supported by the literature).
Ksouda K, Affes H, Atheymen R, Ezzeddine M, Zeghal K, Hammami S. (2014). Autoimmune hepatitis as an adverse effect of long-term methotrexate therapy. Indian J Pharmacol. (53 year old woman with psoriatic arthritis on long term methotrexate therapy [15 mg weekly] with a clinical response and minimal ALT and AST elevations developed fatigue, weight loss and jaundice [bilirubin 12 mg/dL, ALT 620 U/L Alk P 170 U/L, GGT 146 U/L and both ANA and AMA positivity], with resolution of stopping methotrexate and high dose corticosteroid therapy which could eventually be withdrawn).
Hardwick RN, Clarke JD, Lake AD, Canet MJ, Anumol T, Street SM, Merrell MD, et al. (2014). Increased susceptibility to methotrexate-induced toxicity in nonalcoholic steatohepatitis. Toxicol Sci. (Rats given a methionine-choline deficient diet developed steatohepatitis and were more susceptible to hepatic and renal toxicity from high dose methotrexate).
Bath RK, Brar NK, Forouhar FA, Wu GY. (2014). A review of methotrexate-associated hepatotoxicity. J Dig Dis. (Review of the mechanism of action of methotrexate and its hepatotoxicity including clinical features, risk factors, guidelines for monitoring, liver biopsy findings and recommendations for minimizing risk).
Schmajuk G, Miao Y, Yazdany J, Boscardin WJ, Daikh DI, Steinman MA. (2014). Identification of risk factors for elevated transaminases in methotrexate users through an electronic health record. Arthritis Care Res (Hoboken). (Among 659 “users” of methotrexate identified in the electronic health records from the National Veterans Administration Hospital database who were followed for at least 180 days, 126 [19%] had ALT or AST elevations; in multivariate analysis, risk factors for developing abnormalities were obesity, elevated cholesterol levels, baseline liver test abnormalities, use of biologics and no folic acid use).
Strober BE. (2014). Practice gaps. Methotrexate-induced liver toxicity: replacing the liver biopsy. JAMA Dermatol. (Commentary on Lynch et al [2014] mentions that most noninvasive tests such as “Fibrosure”, procollagen III peptide and elastography have unsatisfactory rates of sensitivity and specificity in cross sectional studies; they may perform better when applied prospectively and recommends that “dermatology should abandon the liver biopsy”).
Lynch M, Higgins E, McCormick PA, Kirby B, Nolan N, Rogers S, Lally A, et al. (2014). The use of transient elastography and FibroTest for monitoring hepatotoxicity in patients receiving methotrexate for psoriasis. JAMA Dermatol. (Among 77 adults with psoriasis treated with methotrexate, ultrasound elastography was successful in only 50 [65%] and were abnormally high in 9 [18%], but only one had an elevated ALT level and abnormalities did not correlate with duration of treatment or total dose).
te Loo DM, Hagleitner MM, Coenen MJ. (2014). Is there a role for the MTHFR 677C>T and 1298A>C polymorphisms in methotrexate-induced liver toxicity?. Pharmacogenomics. (Commentary on the possible role of testing for polymorphisms of folate pathway enzymes [MTHFR and DHFR] for their effects on folate metabolism and risk of methotrexate hepatotoxicity, concludes that “it is still unclear”).
Khabbazi A, Kolahi S, Dastgiri S, Hajialiloo M, Nazeri M, Nazeri L, Sheikholeslami Salmasi A, et al. (2014). Safety of less frequent monitoring of liver transaminases levels in rheumatic patients treated with low-dose methotrexate. Int J Rheum Dis. (Among 809 Iranian patients with connective tissue diseases treated with methotrexate for a mean of 32 months who were monitored every 3 months, ALT or AST elevations arose in 108 [13%], leading to dose reduction in 26 [3.2%] and discontinuation in only 4 [0.5%]; no patient developed cirrhosis or end-stage liver disease).
Kubota M, Nakata R, Adachi S, Watanabe K, Heike T, Takeshita Y, Shima M. (2014). Plasma homocysteine, methionine and S-adenosylhomocysteine levels following high-dose methotrexate treatment in pediatric patients with acute lymphoblastic leukemia or Burkitt lymphoma: association with hepatotoxicity. Leuk Lymphoma. (Among 16 children with cancer receiving 26 courses of high dose methotrexate, sequential changes in plasma homocysteine, methionine and S-adenosylhomocysteine levels correlated with concurrent peak elevations in serum ALT [median 28 to 86 U/L] during the 3 days after the infusions).
Park HJ, Park MC, Park YB, Lee SK, Lee SW. (2014). The concomitant use of meloxicam and methotrexate does not clearly increase the risk of silent kidney and liver damages in patients with rheumatoid arthritis. Rheumatol Int. (Among 101 Korean patients with rheumatoid arthritis treated with methotrexate and meloxicam for six months, changes in estimated glomerular filtrate rate and liver stiffness measurements by elastography did not correlate with either the weekly and total doses of either drug).
Hagleitner MM, Coenen MJ, Aplenc R, Patiño-Garcia A, Chiusolo P, Gemmati D, De Mattei M, et al. (2014). The role of the MTHFR 677C>T polymorphism in methotrexate-induced liver toxicity: a meta-analysis in patients with cancer. Pharmacogenomics J. (Among 98 Dutch children receiving high dose methotrexate for acute lymphoblastic leukemia or osteosarcoma, the distribution of 677C >T polymorphisms of the methylene-tetra-hydro-folate reductase gene [MTHFR] showed a trend for a higher rate of hepatotoxicity with TT compared to CC [specific proportions not provided], but the results were considered “indecisive”).
Willner N, Storch S, Tadmor T, Schiff E. (2014). Almost a tragedy: severe methotrexate toxicity in a hemodialysis patient treated for ectopic pregnancy. Eur J Clin Pharmacol. (21 year old woman on long term hemodialysis developed fever, rash and desquamation within 24 hours of receiving intravenous methotrexate [100 mg] for an ectopic pregnancy along with tramadol and dipyrone as analgesics, followed by transient but severe myelosuppression treated with leucovorin rescue; no mention of hepatotoxicity).
Topaloğlu S, Çalık A, Kalaycı O, Çeşmecioğlu E, Çobanoğlu Ü, Uzun Y. (2014). Fibrosing cholestatic hepatitis after methotrexate and prednisone therapy for rheumatoid arthritis. Exp Clin Transplant. (55 year old woman with chronic hepatitis B and rheumatoid arthritis developed worsening liver tests 5 months after starting methotrexate [15 mg/week] and prednisone [10 mg/day] with evidence of HBV reactivation [bilirubin 20 mg/dL, ALT 2272 U/L, HBV DNA > 20 million IU/mL], progressing to hepatic failure despite stopping methotrexate and therapy with lamivudine, and undergoing liver transplantation, the explant demonstrating fibrosing cholestatic hepatitis).
Valentino PL, Church PC, Shah PS, Beyene J, Griffiths AM, Feldman BM, Kamath BM. (2014). Hepatotoxicity caused by methotrexate therapy in children with inflammatory bowel disease: a systematic review and meta-analysis. Inflamm Bowel Dis. (Review of 12 published studies of methotrexate safety, reported 57 of 457 [10.2%] children with inflammatory bowel disease developed varying degrees of biochemical abnormalities which led to discontinuation in approximately half).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, ten were attributed to antineoplastic agents, 6 were due to methotrexate).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases were attributed to antineoplastic agents, 3 of which were due to methotrexate).
Conway R, Low C, Coughlan RJ, O'Donnell MJ, Carey JJ. (2015). Risk of liver injury among methotrexate users: A meta-analysis of randomised controlled trials. Semin Arthritis Rheum. (Metaanalysis of 32 published controlled trials of methotrexate in inflammatory arthridities and inflammatory bowel disease in 13,177 participants found increased rates of minor and major liver enzyme abnormalities with methotrexate compared to comparator arms, but no increased risk of death, cirrhosis or liver failure).
Kim TY, Kim JY, Sohn JH, Lee HS, Bang SY, Kim Y, Kim MY, et al. (2015). Assessment of substantial liver fibrosis by real-time shear wave elastography in methotrexate-treated patients with rheumatoid arthritis. J Ultrasound Med. (Among 185 adults with rheumatoid arthritis being treated with methotrexate, liver stiffness as measured by real-time shear wave elastography was greater than in 81 healthy controls [5.9 vs 5.4 kPa] and was above 8.6 kPa in 9 patients [5%]; liver stiffness did not correlate with total methotrexate dose but did with body mass index).
Schröder T, Schmidt KJ, Olsen V, Möller S, Mackenroth T, Sina C, Lehnert H, et al. (2015). Liver steatosis is a risk factor for hepatotoxicity in patients with inflammatory bowel disease under immunosuppressive treatment. Eur J Gastroenterol Hepatol. (Among 259 patients with inflammatory bowel disease, 73 [28%] had evidence of hepatic steatosis on ultrasound; those with steatosis were older, had higher BMIs and were more likely to have elevated liver tests [29% vs 15%] than those without steatosis but were similar in regards to sex, disease, and immunosuppressive regimen).
Mengual-Moreno E, Lizarzábal-García M, Ruiz-Soler M, Silva-Suarez N, Andrade-Bellido R, Lucena-González M, Bessone F, et al. (2015). Invest Clin. (Among 14 patients with drug induced liver injury seen at a single hospital in Venezuela in 2012-2013, the most common implicated drugs were ibuprofen [n=3], acetaminophen [3], isoniazid [2], and Herbalife products [2]; 1 case was attributed to methotrexate, a 51 year old woman with sarcoidosis treated for 12 months [ALT 214 U/L, Alk P [68 U/L], bilirubin 1.0 mg/dL], resolving with discontinuation).
Osuga T, Ikura Y, Kadota C, Hirano S, Iwai Y, Hayakumo T. (2015). Significance of liver biopsy for the evaluation of methotrexate-induced liver damage in patients with rheumatoid arthritis. Int J Clin Exp Pathol. (Four patients with methotrexate hepatotoxicity who underwent liver biopsy, ages 67 to 80 years on therapy for 3-20 years [ALT 13, 29, 119 and 136 U/L, GGT 16, 14, 32 and 129 U/L, albumin 2.9, 3.0, 4.1 and 4.0 g/dL], liver biopsies not showing cirrhosis in cases 1 and 2 both of whom had ascites, splenomegaly and atrophic liver by CT scan, leading the authors to conclude that “liver biopsy is an unavoidable examination”).
Tsurusawa M, Gosho M, Mori T, Mitsui T, Sunami S, Kobayashi R, Fukano R, et al. (2015). lymphoma committee of the Japanese Pediatric Leukemia/lymphoma Study Group. Statistical analysis of relation between plasma methotrexate concentration and toxicity in high-dose methotrexate therapy of childhood non-Hodgkin lymphoma. Pediatr Blood Cancer. (Among 304 children with non-Hodgkin Lymphoma treated with high doses of methotrexate who had drug levels measured at 24, 48 and 72 hours, rates and severity of renal but not liver and gastrointestinal [GI] toxicities correlated with higher methotrexate levels and rates of liver and GI toxicities were highest with the first and decreased with subsequent courses).
Rabinowich L, Shibolet O. (2015). Drug induced steatohepatitis: An uncommon culprit of a common disease. Biomed Res Int. (Review of the clinical and histologic features of drug induced fatty liver including that caused by aspirin [Reyes], glucocorticoids, iv tetracycline, valproate, alcohol, amiodarone, irinotecan, tamoxifen and methotrexate; mentions that liver enzyme abnormalities develop in 6-24% of patients receiving long term methotrexate but that significant fibrosis or cirrhosis is uncommon [~5%], and end-stage liver disease requiring transplantation is rare [representing 0.07% of liver transplants done in the U.S.]).
Miyagawa K, Shibata M, Noguchi H, Hayashi T, Oe S, Hiura M, Abe S, et al. (2015). Methotrexate-related primary hepatic lymphoma in a patient with rheumatoid arthritis. Intern Med. (56 year old woman with rheumatoid arthritis on methotrexate for six years developed primary large B-cell lymphoma primarily involving the liver [bilirubin 0.7 mg/dL, ALT 23 U/L, Alk P 490 U/L], the tumors responding to stopping methotrexate and six courses of R-CHOP).
Howard SC, McCormick J, Pui CH, Buddington RK, Harvey RD. (2016). Preventing and Managing Toxicities of High-Dose Methotrexate. Oncologist. (Review of toxicities of high doses of methotrexate and their management focusing upon rehydration, urine alkalinization and use of leucovorin doses that reverse the inhibition of intracellular dihydrofolate reductase).
Warren RB, Weatherhead SC, Smith CH, Exton LS, Mohd Mustapa MF, Kirby B, Yesudian PD. (2016). British Association of Dermatologists' guidelines for the safe and effective prescribing of methotrexate for skin disease 2016. Br J Dermatol. (Guidelines for the use of methotrexate in inflammatory skin diseases as well as monitoring for liver injury during therapy recommends routine liver tests and procollagen III peptide levels before and every 3 months during methotrexate therapy, with referral to specialist if levels remain elevated; routine liver biopsy not recommended).
Tang KT, Hung WT, Chen YH, Lin CH, Chen DY. (2016). Methotrexate is not associated with increased liver cirrhosis in a population-based cohort of rheumatoid arthritis patients with chronic hepatitis B. Sci Rep. (Analysis of the Taiwan National Health Insurance Research Database identified 631 incidence cases of rheumatoid arthritis among patients with concurrent chronic hepatitis B, and over an average of 6 years of follow up, the rate of subsequent diagnosis of cirrhosis was the same in those on methotrexate [22 of 358: 6%] as in those who were not [17 of 273: 7%], similarly decompensated cirrhosis arose in 1% of both groups; factors associated with a higher rate of developing cirrhosis were age, male sex and concurrent nonalcoholic fatty liver disease).
Villegas Rubio JA, Cacciavillano W, Rose A, Zubizarreta P, Scopinaro M. (2017). Ambulatory high-dose methotrexate administration in pediatric osteosarcoma patients at a single institution in Argentina. J Pediatr Hematol Oncol. (Over a 4 year period, 150 of 447 courses of high dose methotrexate were given to 24 Argentinian children with osteosarcoma as outpatients, 39% of which were associated with ALT or AST elevations above 5 times ULN, but there were no life threatening events or toxicity related deaths and a total of 324 hospital days were saved).
Humphreys JH, Warner A, Costello R, Lunt M, Verstappen SMM, Dixon WG. (2017). Quantifying the hepatotoxic risk of alcohol consumption in patients with rheumatoid arthritis taking methotrexate. Ann Rheum Dis. (Among 11,839 patients with rheumatoid arthritis receiving methotrexate who were followed in the Clinical Practice Research Datalink, there were 530 episodes of aminotransferase elevations in whom there was a borderline association with 15-21 units of alcohol consumption per week and statistically significant at above 21, suggesting that weekly alcohol intake should be less than 14 per week in persons receiving methotrexate).
Talme T, Nikamo P, Rosenberg P, Ståhle M. (2017). Transient elastography may improve detection of liver fibrosis in psoriasis patients treated with methotrexate. Acta Derm Venereol. (Among 201 patients with psoriasis undergoing transient elastography, mild and severe increase in hepatic stiffness was identified in 38% and 3% on biologics and methotrexate <6 months, 32% and 6% on methotrexate for <24 months and 38% and 9% for >24 months, the major associations with increased stiffness being age, body mass index and diabetes).
Shetty A, Cho W, Alazawi W, Syn WK. (2017). Methotrexate hepatotoxicity and the impact of nonalcoholic fatty liver disease. Am J Med Sci. (Review of the epidemiology, clinical features, histology and natural history of nonalcoholic fatty liver and possible interaction of it with methotrexate hepatotoxicity).
Cabello Zurita C, Grau Pérez M, Hernández Fernández CP, González Quesada A, Valerón Almazán P, Vilar Alejo J, Carretero Hernández G. (2017). Effectiveness and safety of methotrexate in psoriasis: an eight-year experience with 218 patients. J Dermatolog Treat. (Among 218 Spanish patients with psoriasis followed for up to 8 years, 67% received methotrexate as the first systemic treatment, for an average of 17 months, half achieving a clinical response and only 3% stopping therapy because of liver abnormalities, none requiring liver biopsy or developing cirrhosis or end-stage liver disease).
Rongngern P, Chularojanamontri L, Wongpraparut C, Silpa-Archa N, Chotiyaputta W, Pongpaibul A, Charatcharoenwitthaya P. (2017). Diagnostic performance of transient elastography for detection of methotrexate-induced liver injury using Roenigk classification in Asian patients with psoriasis: a retrospective study. Arch Dermatol Res. (Among 41 patients with psoriasis on long term methotrexate [mean 6.4 years] who underwent both liver biopsy and transient elastography [TE] over a 11 year period, 8 had mild [F1, Roenigk stage 3b: TE 4.4-10.0], 2 had moderate fibrosis [F3, Roenigk stage 3a: TE 6.6 and 10], 31 had no fibrosis [Roenigk stage 1: TE 3.4-11.8]; the TE cutoff value for possible fibrosis of 7.1 having a sensitivity of only 50% and specificity of 77%).
Tran-Minh ML, Sousa P, Maillet M, Allez M, Gornet JM. (2017). Hepatic complications induced by immunosuppressants and biologics in inflammatory bowel disease. World J Hepatol. (Review of the liver adverse effects of drugs used to treat inflammatory bowel disease [IBD] mentions that the rate of liver abnormalities in IBD patients receiving methotrexate appears to be low in the range of 5-10% depending upon risk factors such as alcohol intake, obesity, diabetes and concurrent medications as well as use of folic acid; recommends regular monitoring of liver tests and possibly prospective use of transient elastography and other noninvasive means for assessing fibrosis).
Raaby L, Zachariae C, Østensen M, Heickendorff L, Thielsen P, Grønbæk H, Skov L, et al. (2017). Methotrexate use and monitoring in patients with psoriasis: a consensus report based on a Danish expert meeting. Acta Derm Venereol. (A Danish expert meeting on methotrexate monitoring in patients with psoriasis concludes that hepatotoxicity remains a clinical challenge and recommends monitoring with liver enzymes [every 2 weeks for 2 months followed by every 3 months stopping therapy if they are more than 3 fold elevated] and with procollagen III peptide every 6 months [with transient elastography if levels are elevated]).
Ebbesen MS, Nygaard U, Rosthøj S, Sørensen D, Nersting J, Vettenranta K, Wesenberg F, et al. (2017). Hepatotoxicity during maintenance therapy and prognosis in children with acute lymphoblastic leukemia. J Pediatr Hematol Oncol. (Among 385 children with acute lymphoblastic leukemia enrolled in a prospective study of methotrexate and mercaptopurine maintenance therapy, the median ALT values during treatment were 100 U/L, elevations occurring in 91% of children and correlating with mercaptopurine dose and TPMT activity but not with subsequent relapse).
Miele L, Liguori A, Marrone G, Biolato M, Araneo C, Vaccaro FG, Gasbarrini A, et al. (2017). Fatty liver and drugs: the two sides of the same coin. Eur Rev Med Pharmacol Sci. (Review of drugs that can cause fatty liver including methotrexate).
Massart J, Begriche K, Moreau C, Fromenty B. (2017). Role of nonalcoholic fatty liver disease as risk factor for drug-induced hepatotoxicity. J Clin Transl Res. (Extensive review of drug induced liver injury and the role of preexisting obesity and nonalcoholic fatty liver disease [NAFLD] as risk factors and evidence that drugs that cause fatty liver can exacerbate NAFLD).
Tang KT, Chen YM, Chang SN, Lin CH, Chen DY. (2018). Psoriatic patients with chronic viral hepatitis do not have an increased risk of liver cirrhosis despite long-term methotrexate use: Real-world data from a nationwide cohort study in Taiwan. J Am Acad Dermatol. (Analysis of the Taiwan National health Insurance Research Database identified 2417 psoriasis patients with chronic hepatitis B [370 on methotrexate] and 1127 with chronic hepatitis C [174 on methotrexate] who were followed for more than 9 years since the diagnosis and found that the rate of cirrhosis development was the same in those of methotrexate and those who were not: 5% vs 4-5% with hepatitis B and 11% vs 11% with hepatitis C).
Bielen L, Kralj I, Ćurčić E, Vodanović M, Boban A, Božina N. (2018). Acute kidney injury, agranulocytosis, drug-induced liver injury, and posterior reversible encephalopathy syndrome caused by high-dose methotrexate-possible role of low activity ABC and SLC drug transporters. Eur J Clin Pharmacol. (26 year old man with acute lymphoblastic leukemia developed combined bone marrow, renal, hepatic, central nervous system toxicities perhaps due to a heterozygous variant for MTHFR C677T and A1298C as well as coadministration of pantoprazole, ciprofloxacin, piperacillin and ketoprofen).
Shamberg L, Vaziri H. (2018). Hepatotoxicity of inflammatory bowel disease medications. J Clin Gastroenterol. (Review of drugs for inflammatory bowel disease and their potential for hepatotoxicity mentions that rates of serum enzyme elevations with methotrexate therapy is lower in IBD than in rheumatic diseases).
Ortega-Alonso A, Andrade RJ. (2018). Chronic liver injury induced by drugs and toxins. J Dig Dis. (Review of the frequency, course and causes of chronic liver injury from medications, rates of which have varied from 6-39% depending upon definition, clinical patterns being steatohepatitis [as with methotrexate], nodular regenerative hyperplasia and cirrhosis [possibly with methotrexate], autoimmune hepatitis [reported with methotrexate] and vanishing bile duct syndrome [usually due to severe acute cholestatic hepatitis]).
Mori S, Arima N, Ito M, Fujiyama S, Kamo Y, Ueki Y. (2018). Non-alcoholic steatohepatitis-like pattern in liver biopsy of rheumatoid arthritis patients with persistent transaminitis during low-dose methotrexate treatment. PLoS One. (Among 846 Japanese patients with rheumatoid arthritis on methotrexate therapy monitored for 1 year, 51 had persistent ALT or AST elevations and were on average older, more like to be obese, to have diabetes, and elevated cholesterol and uric acid levels, but had similar total methotrexate dose and duration of treatment to those without elevations; ultrasonography showing increased hepatic fat in 42 while liver biopsy in 32 showed steatosis, 22 with NASH- like changes, 15 with advanced fibrosis but none with cirrhosis).
Svanström H, Lund M, Melbye M, Pasternak B. (2018). Concomitant use of low-dose methotrexate and NSAIDs and the risk of serious adverse events among patients with rheumatoid arthritis. Pharmacoepidemiol Drug Saf. (Analysis of 17,200 new users of low dose methotrexate from the Danish National Patient Register found an increased risk of serious adverse events among those taking an NSAID concurrently compared to those on methotrexate alone; rates per 1000 person-years being 12.1 vs 11.0, rates of renal and hematologic adverse events being higher but hepatotoxicity rates being lower [0.3 vs 0.6 per 1000 person-years]).
Hakamata J, Hashiguchi M, Kaneko Y, Yamaoka K, Shimizu M, Maruyama J, Takeuchi T, et al. (2018). Risk factors for abnormal hepatic enzyme elevation by methotrexate treatment in patients with rheumatoid arthritis: A hospital based-cohort study. Mod Rheumatol. (Among 114 Japanese patients with rheumatoid arthritis starting treatment with methotrexate and monitored for one year, 32 developed liver enzyme elevations [28%], rates being higher in those with in those with genetic polymorphisms of ABCB1 3435C>T [34% vs 16%] but not for rates of elevations >2 times ULN [14% vs 14%]).
Cheng HS, Rademaker M. (2018). Monitoring methotrexate-induced liver fibrosis in patients with psoriasis: utility of transient elastography. Psoriasis (Auckl). (Review of issues of monitoring patients with psoriasis on methotrexate therapy, recommending use of transient elastography at baseline and every three years if stiffness measurements are <7.5, yearly if 7.5-9.5, stopping therapy or further investigations and possibly liver biopsy if >9.5).
Fiore M, Leone S, Maraolo AE, Berti E, Damiani G. (2018). Liver Illness and Psoriatic Patients. Biomed Res Int. (Review of liver complications of psoriasis and its therapy discusses methotrexate hepatotoxicity which may be more frequent in patients with psoriasis than in those with rheumatoid arthritis or inflammatory bowel disease).
Wood PR, Caplan L. (2018). Drug-induced gastrointestinal and hepatic disease associated with biologics and nonbiologic disease-modifying antirheumatic drugs. Rheum Dis Clin North Am. (Review of drug induced gastrointestinal and liver injury due to disease modifying antirheumatic drugs including methotrexate, azathioprine, tofacitinib, sulfasalazine, hydroxychloroquine and leflunomide as well as biologics such as tocilizumab, ustekinumab and infliximab).
(2018). Drugs for inflammatory bowel disease. Med Lett Drugs Ther. (Concise review of the management of inflammatory bowel disease and safety and efficacy of drugs used, includes mention of methotrexate as an alternative to azathioprine and mercaptopurine, its adverse events including hepatotoxicity).
Efe C, Ozaslan E, Purnak T. (2018). Methotrexate in the treatment of autoimmune hepatitis. Clin Gastroenterol Hepatol. (37 year old woman developed autoimmune hepatitis that was satisfactorily controlled with prednisolone and azathioprine, later developing rheumatoid arthritis and switched to methotrexate which controlled both the arthritis and the hepatitis, serum aminotransferase levels remaining normal).
Haridy J, Nicoll A, Sood S. (2018). Methotrexate therapy for autoimmune hepatitis. Clin Gastroenterol Hepatol. (Among 11 Australian patients with refractory autoimmune hepatitis and lack of response or intolerance to azathioprine, switching to methotrexate [7.5-20 mg/wk] lead to a complete biochemical remission in 6 who had a long term response, but was associated with worsening of the hepatitis in the remaining 5 which led to discontinuation of methotrexate).
Alfaro-Lara R, Espinosa-Ortega HF, Arce-Salinas CA, PRECIS study group. (2019). all physicians belong to Division of Internal Medicine. Hospital Central Sur de Pemex. Systematic review and meta-analysis of the efficacy and safety of leflunomide and methotrexate in the treatment of rheumatoid arthritis. Reumatol Clin. (Systematic review of 6 publications on efficacy and safety of leflunomide vs methotrexate indicated that leflunomide was probably as effective as methotrexate, and was less likely to cause serum aminotransferase elevations [6.3% vs 15%]).
Miyata M, Kuroda M, Unakami M, Tasaki K, Migita K, Ohira H. (2019). Validation of the fibrosis-4 (FIB-4) index in the diagnosis of liver disease of rheumatoid arthritis patients treated with methotrexate. Mod Rheumatol. (Fib-4 scores were calculated on 395 patients with rheumatoid arthritis on long term methotrexate therapy focusing on 14 who underwent liver biopsy for suspect hepatotoxicity among whom Fib-4 scores improved after stopping therapy).
Karlsson Sundbaum J, Eriksson N, Hallberg P, Lehto N, Wadelius M, Baecklund E. (2019). Methotrexate treatment in rheumatoid arthritis and elevated liver enzymes: A long-term follow-up of predictors, surveillance, and outcome in clinical practice. Int J Rheum Dis. (Among 213 patients with rheumatoid arthritis started on methotrexate and followed for an average of 4.3 years with regular monitoring, 44 [21%] developed ALT elevations and 7 [3%] stopped therapy because of persistent elevations, most of whom had elevations during follow up off of methotrexate, but no patients develop cirrhosis or signs hepatic failure).
Pivovarov K, Zipursky JS. (2019). Low-dose methotrexate toxicity. CMAJ. (Recommendations on use of low dose methotrexate in rheumatoid arthritis, inflammatory arthritidies and Crohn disease advises measuring routine liver tests liver tests before starting, followed by monitoring every 2-4 weeks for the first 3 months, every 8-12 weeks for the second 3 months and every 12 weeks thereafter, and taking folic acid [1 mg] on days that methotrexate is not taken).
Labadie JG, Jain M. (2019). Noninvasive tests to monitor methotrexate-induced liver injury. Clin Liver Dis (Hoboken). (Brief review of noninvasive tests of fibrosis that can be used to monitor for methotrexate hepatotoxicity including transient elastography, procollagen III peptide and Fibrosure).
Lertnawapan R, Chonprasertsuk S, Siramolpiwat S. (2019). Association between cumulative methotrexate dose, non-invasive scoring system and hepatic fibrosis detected by Fibroscan in rheumatoid arthritis patients receiving methotrexate. Int J Rheum Dis. (Among 108 patients with rheumatoid arthritis treated with low dose methotrexate who underwent transient elastography, 29 had elevations in liver stiffness measurements [kPa >7] and had significantly higher average BMI, longer duration of therapy and total methotrexate dose, and higher ALT, GGT and INR levels than those with normal liver stiffness; but were similar in age, gender, alcohol and concurrent medication use, levels of HbA1c, creatinine and cholesterol, and scores for APRI and Fib-4).
Allard J, Le Guillou D, Begriche K, Fromenty B. (2019). Drug-induced liver injury in obesity and nonalcoholic fatty liver disease. Adv Pharmacol. (Summary of clinical and histologic features of drug induced liver injury in patients with obesity and nonalcoholic fatty liver disease (NAFLD), methotrexate having similar clinical and histologic features with NAFLD and hepatotoxicity seemingly more common in obese patients and those with underlying NAFLD).
García DS, Saturansky EI, Poncino D, Martínez-Artola Y, Rosenberg S, Abritta G, Ascimani-Peña C, Cravero A. (2019). Hepatic toxicity by methotrexate with weekly single doses associated with folic acid in rheumatoid and psoriatic arthritis. what is its real frequency?. Ann Hepatol. (Application of the Roussel Uclaf Causality Assessment Method to 5 patients with psoriatic arthritis who developed ALT elevations during therapy suggested that all 5 were “improbable”, 3 being more likely due to concurrent use of NSAIDs and 2 being more likely due to nonalcoholic fatty liver).
Kelgeri C, Ramakrishna SH, Brown RM, Al-Abadi E, Gupte GL. (2019). Liver injury in children with long-term low-dose methotrexate. Acta Paediatr. (Among 742 children on long term methotrexate for nonmalignant disease, 14 underwent liver biopsy to guide therapy, 12 of whom were advised to continue or restart methotrexate and the two who stopped therapy had moderate-to-severe fibrosis and both had subsequent normalization of serum enzyme elevations).

## OTHER REFERENCE LINKS

1 Recent References on Methotrexate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Methotrexate/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Methotrexate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Methotrexate)